# Protease Inhibitors (HIV)

## OVERVIEW

The human immunodeficiency virus (HIV) protease inhibitors are a broad class of agents that are widely used in the therapy and prevention of HIV infection and the acquired immunodeficiency syndrome (AIDS). All of the currently available protease inhibitors have been associated with transient and usually asymptomatic elevations in serum aminotransferase levels, and several (atazanavir, indinavir) with mild-to-moderate elevations in indirect and total bilirubin concentration. The protease inhibitors are rare causes of clinically apparent, acute liver injury. In HBV or HCV coinfected patients, antiretroviral therapy with highly active antiretroviral therapy (HAART) including protease inhibitors may result in an exacerbation of the underlying chronic hepatitis B or C.

The antiretroviral protease inhibitors act by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Most of these agents were developed by rational drug design based upon chemical structures that would interact with the catalytic site of the HIV protease, based upon x-ray crystallographic studies defining the three-dimensional molecular structure of the protease. For these reasons, the protease inhibitors are heterogeneous molecules with little structural similarity, most of which are peptide-like and resemble the short peptide that is cleaved by the viral protease (usually the N terminal side of the middle proline residue is phenylalanine-proline-proline).

The initial HIV protease approved for use in the United States was ritonavir (1996), followed in short order by indinavir (1996), nelfinavir (1997), saquinavir (1997), amprenavir (1999), lopinavir/ritonavir (2000), atazanavir (2003), fosamprenavir (2003), tipranavir (2005), and darunivir (2006). The potencies of these agents are similar and the major reason for using one or the other relates to pharmacokinetics (whether they are taken once vs multiple times daily), tolerance and presence of antiviral resistance.

Most of the HIV protease inhibitors are metabolized by the liver, via the cytochrome P450 drug metabolizing enzymes. Importantly, all of the approved HIV protease inhibitors have the potential for significant drug-drug interactions because of their potential in inhibiting drug metabolizing enzymes, most commonly CYP 3A4. Ritonavir is the most potent CYP 3A4 inhibitor and, for this reason, is often combined in low doses (100 to 200 mg daily) with other protease inhibitors to produce a "booster" effect, increasing the plasma levels and half-life of the protease inhibitor without significantly increasing side effects. Cobicistat is a more recently introduced pharmacological enhancer which has inhibitory activity against several drug metabolizing enzymes besides CYP 3A4, including CYP 2D6 and the P-glycoprotein transporter, which makes it a potent means of increasing drug levels of agents metabolized by the cytochrome P450 system. Several fixed combinations of cobicistat with antiretroviral agents have been approved for use in the United States, including combinations with atazanavir (Evotaz), elvitegravir (Genvoya and Stribild), and darunavir (Prezcobix). Cobicistat is also available as a separate oral tablet of 150 mg (Tybos).

As with other antiretroviral agents, therapy with the protease inhibitors is limited by the development of antiviral resistance. For this reason, the protease inhibitors are given in combination with other antiretroviral agents, belonging to other drug classes, such as the nucleoside analogues, the nonnucleoside reverse transcriptase inhibitors and the miscellaneous agents. Introduction of the HIV protease inhibitors into clinical practice was followed by a dramatic increase in survival in HIV-infected populations, a major accomplishment towards the goal of decreasing the burden of HIV infection.

The protease inhibitors are associated with four main forms of hepatotoxicity. First, are the mild-to-moderate elevations in serum aminotransferase and alkaline phosphatase levels that occur in a high proportion of patients taking protease inhibitor-containing antiretroviral regimens. Moderate-to-severe elevations in serum aminotransferase levels (above 5 times the upper limit of normal) are found in 2% to 18% of patients depending upon the agent, the frequency of monitoring and, most importantly, the presence of HBV or HCV coinfection. In patients with HIV without HCV or HBV infection ("mono-infection"), ALT and AST elevations are less frequent and levels above 5 times the upper limit of normal are reported in only 1% to 4% of recipients. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Outside of carefully monitored clinical trials, serum enzyme elevations are an uncommon reason for discontinuing therapy.

A second liver related reaction to protease inihibitor therapy is hyperbilirubinemia without other evidence of liver injury. Therapy with two protease inhibitors–indinavir and atazanavir–is associated with elevations in unconjugated (indirect) and total serum bilirubin, and can cause clinically apparent jaundice in up to 10% of patients. These elevations are due to the inhibition of UDP glucuronyl transferase, the hepatic enzyme responsible for conjugation of bilirubin that is deficient in Gilbert syndrome. The hyperbilirubinemia is usually mild, averaging 0.9-1.5 mg/dL, but can be more marked in patients with Gilbert syndrome with increases of 2.5 mg/dL or more and clinical jaundice. The jaundice, however, is not indicative of hepatic injury. Nevertheless, the jaundice caused by these agents can be distressing to the patient and is an occasional reason for discontinuation.

A third pattern of hepatotoxicity attributed to protease inhibitors is idiosyncratic, clinically apparent acute liver injury which has been reported with most agents but is decidedly rare. The few cases that have been reported have usually arisen within 1 to 12 weeks of starting therapy and the pattern of serum enzyme elevations has varied from hepatocellular to mixed to cholestatic. Signs of allergy or hypersensitivity (fever, rash, eosinophilia) can occur but are rare, as is autoantibody formation. The acute liver injury due to the protease inhibitors is usually self-limited, but it can be severe, and isolated cases of acute liver failure have been reported particularly in patients with preexisting, underlying liver disease.

Finally, the fourth pattern of hepatotoxicity that occurs during protease inhibitor therapy is the exacerbation of an underlying chronic hepatitis B or C in coinfected individuals started on highly active antiretroviral therapy. The flare of hepatitis typically arises 2 to 12 months after starting therapy and is associated with a hepatocellular pattern of serum enzyme elevations and increases (followed by falls) in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. These flares can be severe and fatal instances have been reported with many of the protease inhibitors.

The protease inhibitors have not been linked to lactic acidosis and acute fatty liver that are associated with several nucleoside analogue reverse transcriptase inhibitors such as stavudine, didanosine and zidovudine, and rare cases of acute hypersensitivity associated hepatotoxicity as occurs with nevirapine, efaverenz and abacavir. However, because the protease inhibitors are usually given in combination with several other antiretroviral medications, identification of the drug causing the hepatic injury can be difficult.

Each of the following HIV protease inhibitors are discussed individually, but the references are combined and given below.

- Amprenavir
- Atazanavir
- Darunavir
- Fosamprenavir
- Indinavir
- Lopinavir
- Nelfinavir
- Ritonavir
- Saquinavir
- Tipranavir

## ANNOTATED BIBLIOGRAPHY

References updated: 01 September 2017

Abbreviations used: HIV, human immunodeficiency virus; HCV, hepatitis C virus; HBV, hepatitis B virus; ULN, upper limit of normal; /r, agent boosted with ritonavir; /c, agent boosted with cobicistat.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents mentions that risk of liver injury with different protease inhibitors is controversial, but that tipranavir, darunavir, lopinarivr and ritonavir are the leading causes in most case reports and reviews on the topic).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Freiman JP, Helfert KE, Hammrell MR, Stein DS. Hepatomegaly with severe steatosis in HIV-seropositive patients. AIDS 1993; 7: 379-85. (8 patients with HIV who developed severe hepatomegaly and marked steatosis which was associated with hepatic failure and lactic acidosis, 6 being fatal and 2 with recovery; all had received zidovudine, but for varying periods and often stopped well before onset of symptoms from hepatotoxicity). 8471200
Styrt B, Freiman JP. Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am 1995; 24: 839-52. (Review of liver toxicity of antiviral agents, before availability of protease inhibitors). 8749901
Bräu N, Leaf HL, Wieczorek RL, Margolis DM. Severe hepatitis in three AIDS patients treated with indinavir. Lancet 1997; 349: 924-5. (2 men and 1 woman, ages 37-52 years, developed abdominal pain followed by jaundice 4-10 days after adding indinavir to an antiretroviral regimen [peak bilirubin 17.5, 6.1 and 2.5 mg/dL, ALT 690, 1602 and 1875 U/L, Alk P 145, 49 and 159 U/L]; 1 patient with HBsAg died, the 2 others [one with HCV] resolved on stopping indinavir). 9093260
Matsuda J, Gohchi K. Severe hepatitis in patients with AIDS and haemophilia B treated with indinavir. Lancet 1997; 350: 364. (27 year old man with hemophilia B and HCV [maximal ALT 94 U/L] had worsening ALT levels [60 rising to 807 U/L] and eosinophilia 6 months after adding indinavir to an antiretroviral regimen, and was maintained on indinavir with persistence of ALT elevations [187 U/L]). 9251655
Carr A, Cooper DA. Restoration of immunity to chronic hepatitis B infection in HIV-infected patient on protease inhibitor. Lancet 1997; 349: 995-6. (34 year old with HIV-HBV coinfection developed rise in ALT levels [80 to 310 to 680 U/L] 5 weeks after starting ritonavir, with subsequent worsening before clearance of both HBeAg and HBV DNA followed by fall of ALT into the normal range; interpreted as HBeAg seroconversion possibly triggered by immune constitution). 9100629
Carr A, Brown D, Cooper DA. Portal vein thrombosis in patients receiving indinavir, an HIV protease inhibitor. AIDS 1997; 11: 165-8. (Two patients presenting with portal hypertension without cirrhosis while on antiretroviral therapy with indinavir and stavudine, found to have evidence of portal vein thrombosis, but other possibility was nodular regenerative hyperplasia). 9365776
Hammer SM, Squires KE, Hughes MD, Grimes JM, Demeter LM, Currier JS, Eron JJ Jr, et al. A controlled trial of two nucleoside analogues plus indinavir in persons with human immunodeficiency virus infection and CD4 cell counts of 200 per cubic millimeter or less. AIDS Clinical Trials Group 320 Study Team. N Engl J Med 1997; 337: 725-33. (Controlled trial of indinavir with 2 nucleoside analogues or the 2 nucleosides alone in 1156 patients with HIV infection; no mention of hepatotoxicity or ALT elevations). 9287227
Vandercam B, Moreau M, Horsmans C, Gala JL. Acute hepatitis in a patient treated with saquinavir and ritonavir: absence of cross-toxicity with indinavir. Infection 1998; 26: 313. (46 year old man with HIV infection developed nausea within hours of starting stavudine, saquinavir and ritonavir, recurring on restarting [bilirubin normal, ALT 1833 U/L, GGT 175 U/L, no eosinophilia], resolving rapidly and not recurring on starting stavudine, lamivudine and indinavir). 9795794
Vergis E, Paterson DL, Singh N. Indinavir-associated hepatitis in patients with advanced HIV infection. Int J STD AIDS 1998; 9: 53. (46 year old man with HIV infection developed pain and jaundice 46 days after adding indinavir to antiretroviral regimen [bilirubin 3.7 rising to 12.2 mg/dL, ALT 123 U/L, Alk P 136 U/L], followed by ascites and coagulopathy; biopsy showed fat and necrosis, ultimately resolving: Case 1, indinavir). 9518018
Vento S, Garofano T, Renzini C, Casali F, Ferraro T, Concia E. Enhancement of hepatitis C virus replication and liver damage in HIV-coinfected patients on antiretroviral combination therapy. AIDS 1998; 12: 116-7. (Among 51 patients with HIV-HCV coinfection started on highly active antiretroviral therapy, rises in HCV RNA levels at one month with worsening of ALT, falls in HIV RNA levels and rises in CD4 count were common; while liver biopsy in 31 patients showed worsening and 7 had clinical decompensation). 9456265
Arribas JR, Ibanez C, Ruiz-Antoran B, Pena JM, Esteban-Calvo C, Frias J, Vazquez JJ, et al. Acute hepatitis in HIV-infected patients during ritonavir treatment. AIDS 1998; 12: 1722-4. (Among 141 patients treated with full dose ritonavir, 10 developed hepatitis [9 with HCV coinfection] arising within 2 months of starting, 7 with symptoms and 6 with jaundice [bilirubin 0.8 to 16 mg/dL, ALT 418 to 1206 U/L], all resolving, two without dose modification). 9764797
Rodiguez-Rosado R, Garcia-Samaniego J, Soriano V. Hepatotoxicity after introduction of highly active antiretroviral therapy. AIDS 1998; 12: 1256. (Analysis of first 187 patients starting highly active antiretroviral therapy; rise in ALT >2 times baseline occurred in 14%, bilirubin >2.5 mg/dL in 4%; 4 patients developed hepatic decompensation and one died). 9677182
Mina J, Flexman J, French MA. Hepatitis C virus-associated hepatitis following treatment of HIV-infected patients with HIV protease inhibitors: an immune restoration disease? AIDS 1998; 12: 2289-93. (Analysis of course of 3 of 133 patients on antiretroviral therapy who developed acute liver injury; all had HCV infection and hepatitis appeared with immune restoration, often with development of anti-HCV in a patient with long standing HCV RNA positivity). 9863871
Karras A, Rabian C, Zylberberg H, Hermine O, Duchatelle V, Durand F, Valla D, et al. Severe anoxic necrosis in an HIV-1-hepatitis C virus-co-infected patient starting antiretroviral triple combination therapy. AIDS 1998; 12: 827-9. (30 year old man with HIV-HCV coinfection developed red cell aplasia and severe anemia [hemoglobin 3 g/dL] 2 months after starting lamivudine, zidovudine and indinavir, with acute abdominal pain [bilirubin 12.7 mg/dL, ALT 35 times ULN, Alk P normal], recovering in 2 weeks of stopping and tolerating restarting lamivudine, zalcitabine and indinavir without recurrence; biopsy showed ischemic hepatitis). 9619823
Picard O, Rosmorduc O, Cabane J. Hepatotoxicity associated with ritonavir. Ann Intern Med 1998; 129: 670-2. (28 year old woman with HIV infection developed elevated ALT [133 U/L] 5 weeks after adding ritonavir and stavudine to lamivudine with rapid resolution, but recurrence 5 weeks after restarting with abdominal pain, jaundice, hepatic failure and lactic acidosis [bilirubin 19.4 mg/dL, ALT 254 U/L, prothrombin index 22%], resolving slowly within 8 weeks of stopping; later tolerated lamivudine and stavudine alone). 9786823
Havlir DV, Lange JM. New antiretrovirals and new combinations. AIDS 1998; 12 Suppl A: S165-74. (Review of new agents for HIV infection, including nelfinavir, nevirapine, delaviridine, efavirenz and abacavir; most significant toxicities discussed include diarrhea for nelfinavir, rash and hepatitis for nevirapine, rash for delavirdine; little information available on toxicities of other agents). 9632999
Rutschmann OT, Negro F, Hirschel B, Hadengue A, Anwar D, Perrin LH. Impact of treatment with human immunodeficiency virus (HIV) protease inhibitors on hepatitis C viremia in patients coinfected with HIV. J Infect Dis 1998; 177: 783-5. (Analysis of HCV RNA levels in 19 patients with HIV-HCV coinfection; after 6 weeks of highly active antiretroviral therapy, HCV RNA levels increased slightly [mean = +0.4 log IU/mL], returning to baseline by 4 months with little or no change in ALT levels). 9498464
Zylberberg H, Chaix ML, Rabian C, Rouzioux C, Aulong B, Bréchot C, Viard JP, et al. Tritherapy for human immunodeficiency virus does not modify replication of hepatitis C virus in coinfected subjects. Clin Infect Dis 1998; 26:1104-6. (Among 22 patients with HIV-HCV coinfection started on various regimens of highly active antiretroviral therapy, HIV levels decreased and CD4 counts increased, but ALT and HCV RNA levels did not change significantly). 9597236
Zylberberg H, Pialoux G, Carnot F, Landau A, Bréchot C, Pol S. Rapidly evolving hepatitis C virus-related cirrhosis in a human immunodeficiency virus-infected patient receiving triple antiretroviral therapy. Clin Infect Dis 1998; 27:1255-8. (36 year old with HIV-HCV coinfection developed ascites 9 months after starting lamivudine, indinavir and stavudine [bilirubin 2.1 mg/dL, ALT 60 U/L, and Alk P 107 U/L], with subsequent liver failure; biopsy showed nodularity and "cirrhosis"). 9827279
Rockstroh JK, Theisen A, Kaiser R, Sauerbruch T, Spengler U. Antiretroviral triple therapy decreases HIV viral load but does not alter hepatitis C virus (HCV) serum levels in HIV-HCV-co-infected haemophiliacs. AIDS 1998; 12: 829-30. (Prospective study of 26 patients with hemophilia and HIV-HCV coinfection started on saquinavir or indinavir on top of chronic therapy with two nucleoside analogues; despite improvements in CD4 counts and HIV RNA levels at 3 months, HCV RNA and ALT levels did not change). 9619824
Mastroianni C, Trinhieri V, Santopadre P, Lichtner M, Forcina G, D'Agostino C, Corpolongo A, et al. Acute clinical hepatitis in an HIV-seropositive hepatitis B carrier receiving protease inhibitor therapy. AIDS 1998; 12: 1939-40. (62 year old man with HIV-HBV coinfection with normal ALT and no HBeAg developed abdominal pain 12 weeks after starting lamivudine, stavudine and ritonavir [ALT 1340 U/L and presence of HBeAg, HBV DNA and IgM anti-HBc indicative of reactivation], resolving in 8 weeks of stopping despite persistence of HBeAg). 9792403
Pai V, Nahata M. Nelfinavir mesylate: a protease inhibitor. Ann Pharmacother 1999; 33: 325-39. (Review of the structure, activity, pharmacology, safety and tolerance of nelfinavir, an antiretroviral agent developed using rational drug design as an agent that binds to active site of HIV-1 protease blocking its activity; most common side effects are diarrhea [14-32%], nausea [2-7%] and skin rash [3-4%]; ALT elevations in 1-3%, and lipodystrophy with long term use; also a competitive inhibitor of CYP 3A4 and has major drug-drug interactions). 10200859
Orenstein R, LeGall-Salmon E. HIV treatment-associated hepatitis. AIDS Read 1999; 9: 339-46. (Review of antiretrovirals and liver injury; by 1998, 80% of antiretroviral regimens included a protease inhibitor; ritonavir most commonly associated with liver injury, with several instances of acute hepatitis arising within 12-82 days, resolving in 1-2 months, 2 positive rechallenges; cases also reported with indinavir, less know about saquinavir and amprenavir). 12737123
Velasco M, Moran A, Teliez MJ. Resolution of chronic hepatitis B after ritonavir treatment in an HIV-infected patient. N Engl J Med 1999; 340: 1765-6. (35 year old with HIV-HBV coinfection developed nausea 9 weeks after adding ritonavir to didanosine and zidovudine [ALT 503 U/L], resolving despite continuing antiretrovirals, ultimately clearing HBV DNA and HBsAg). 10357637
Nigro I, Romano F, Tosto S, Zagami A, Bruno S, Nunnari A. Severe hepatitis in an HIV-positive subject under treatment with a protease inhibitor. Ital J Gastroenterol 1999; 31: 85-6. (37 year old man with HIV-HBV coinfection, developed jaundice 20 days after adding indinavir to zidovudine and zalcitabine [bilirubin 11.2 mg/dL, ALT 1608 U/L, borderline IgM anti-HBc, CD4 cells having risen from 4 to 97], resolving within 7 weeks of stopping with clearance of HBsAg; anti-HCV was also present, but HCV RNA testing was not done). 10091111
Ragni MV, Bontempo FA. Increase in hepatitis C virus load in haemophiliacs during treatment with highly active antiretroviral therapy. J Infect Dis 1999; 180: 2027-9. (Analysis of 21 patients with hemophilia and HIV-HCV coinfection starting highly active antiretroviral therapy; HCV RNA levels tended to increase with prolonged therapy [48 weeks], one developed decompensation). 10558963
Benveniste O, Longuet P, Duval X, Le Moing V, Leport C, Vildé JL. Two episodes of acute renal failure, rhabdomyolysis, and severe hepatitis in an AIDS patient successively treated with ritonavir and indinavir. Clin Infect Dis 1999; 28: 1180-1. (34 year old man with HIV-HCV coinfection developed fever and jaundice 6 days after starting ritonavir [bilirubin 12.3 mg/dL, ALT 491 U/L, creatinine 4.1 mg/dL], resolving with stopping and then tolerating indinavir, stavudine and lamivudine for 1 year when presented with lactic acidosis and jaundice [bilirubin 10.2 mg/dL, ALT 234 U/L, CPK 3074 U/L], resolving with stopping; unclear which agent[s] were responsible for second episode). 10452668
Savès M, Raffi F, Clevenbergh P, Marchou B, Waldner-Combernoux A, Morlat P, Le Moing V, et al., The APROCO Study Group. Hepatitis B or C virus infection is a risk factor for severe hepatic cytolysis after initiation of a protease inhibitor-containing antiretroviral regimen in human immunodeficiency virus-infected patients. Antimicrob Agents Chemother 2000; 44: 3451-5. (Among 1047 patients with HIV infection who were started on protease inhibitors, ALT elevations >5 times ULN occurred in 5 per patient-year, HCV infection raised the risk 8-fold and HBsAg 6.7-fold, but rate did not differ by specific protease inhibitor used). 11083658
Pai V, Koranyi K, Nahata M. Acute hepatitis and bleeding possibly induced by zidovudine and ritonavir in an infant with HIV infection. Pharmacotherapy 2000; 20: 1135-40. (9 year old boy with HIV infection and multiple complications developed fever, thrombocytopenia and hepatitis 2 months after starting zidovudine, lamivudine and ritonavir with progressive liver failure and severe bleeding after liver biopsy; difficult to assign specific causality). 10999509
Carr A, Miller J, Law M, Cooper DA. A syndrome of lipoatrophy, lactic acidemia and liver dysfunction associated with HIV nucleoside analogue therapy: contribution to protease inhibitor related syndrome. AIDS 2000; 18: F25-32. (Description of 14 patients with lipodystrophy and liver dysfunction who were never treated with protease inhibitors, most having received stavudine [86%] or didanosine [71%] for more than 6 months and most developing hyperlactatemia, ALT elevations and symptoms of weight loss, nausea and fatigue; most recovered slowly upon withdrawal). 10716495
Puoti M, Gargiulo F, Roldan EQ, Chiodera A, Palvarini L, Spinetti A, Zaltron S, et al. Liver damage and kinetics of hepatitis C virus and human immunodeficiency virus replication during the early phases of combination antiretroviral treatment. J Infect Dis 2000; 181: 2033-6. (Monitoring viral levels during initiation of antiretroviral therapy with either nevirapine or indinavir with lamivudine and stavudine in 12 patients with HIV and HCV coinfection found slight rise in HCV RNA during weeks 1-3 of therapy, with no consistent change in ALT). 10837187
Puoti M, Spinetti A, Ghezzi A, Donato F, Zaltron S, Putzolu V, Quiros-Roldan E, et al., Hepatitis-HIV Study Group. Mortality for liver disease in patients with HIV infection: a cohort study. J Acquir Immune Defic Syndr 2000; 24: 211-7. (Analysis of 308 in hospital deaths in patients with AIDS between 1987-1995, found 35 who died of liver failure [12%]; risk factors were hepatitis B and alcohol abuse; HCV and HDV were significant in univariate analysis, but antiretroviral use was not). 10969344
Gisolf E, Dreezen C, Danner S, Weel JL, Weverling GJ. Prometheus Study Group. Risk factors for hepatotoxicity in HIV-1 infected patients receiving ritonavir and saquinavir with or without stavudine. Clin Infect Dis 2000; 3: 1234-9. (Among 218 patients with HIV infection starting antiretroviral therapy, 18 [9%] developed liver enzyme elevations at an average of 12 weeks [ALT 150 rising to 1890 U/L]; risk factors were HBV coinfection and stavudine use). 11073757
den Brinker M, Wit FW, Wertheim-van Dillen PM, Jurriaans S, Weel J, van Leeuwen R, Pakker NG, et al. Hepatitis B and C virus co-infection and the risk for hepatotoxicity of highly active antiretroviral therapy in HIV-1 infection. AIDS 2000; 14: 2895-902. (Retrospective analysis of 394 HIV infected patients starting antiretroviral therapy; liver enzyme elevations occurred in 45% with HBV, 33% with HCV, and 12% with neither, onset averaging 25 weeks after starting; HBeAg loss in 7 patients). 11153671
Reijers MH, Weigel HM, Hart AA, Ten Kate RW, Mulder JW, Reiss P, Schultemaker H, et al. Toxicity and drug exposure in a quadruple drug regimen in HIV-1 infected patients participating in the ADAM study. AIDS 2000; 14: 59-68. . (Among 65 treatment-naïve patients starting stavudine, lamivudine, nelfinavir or saquinavir, 12 had liver enzyme elevations that required discontinuation, but this did not correlate with excessively high drug levels). 10714568
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA 2000; 283: 74-80. (Among 298 patients with HIV infection, ALT elevations >5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection). 10632283
Velasco M, Guijarro C. Elevated liver enzymes following initiation of antiretroviral therapy. JAMA 2000; 283: 2526-7. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C which may be misdiagnosed as hepatotoxicity). 10815112
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Elevated liver enzymes following initiation of antiretroviral therapy JAMA 2000; 283: 2526-7. (Reply to Velasco and Guijarro pointing out that the majority of the ALT elevations described could not be attributed to immune reconstitution). 10815113
Melvin DC, Lee JK, Belsey E, Arnold J, Murphy RL. The impact of co-infection with hepatitis C virus and HIV on the tolerability of antiretroviral therapy. AIDS 2000; 14: 463. (The rate of discontinuation of antiretroviral therapy for hepatotoxicity was 17% among 45 HIV-HCV coinfected patients compared to only 6.8% of 50 matched HIV monoinfected patients). 10770552
Gavazzi G, Bouchard O, Leclercq P, Morel-Baccard C, Bosseray A, Dutertre N, Micoud M, et al. Change in transaminases in hepatitis C virus- and HIV-coinfected patients after highly active antiretroviral therapy: differences between complete and partial virologic responders? AIDS Res Hum Retroviruses 2000 20; 16: 1021-3. (Prospective study of 22 patients with HIV-HCV coinfection starting highly active antiretroviral therapy; levels of HIV fell, CD4 counts rose, but HCV RNA levels did not change between baseline and month 12 both in responders and nonresponders to antiretroviral therapy). 10933615
Zucker SD, Qin X, Rouster SD, Yu F, Green RM, Keshavan P, Feinberg J, et al. Mechanism of indinavir-induced hyperbilirubinemia. Proc Natl Acad Sci U S A 2001; 98: 12671-6. (Analysis of effects of indinavir on UDP glucuronyltransferase activity in vitro and in vivo, showing competitive inhibition by indinavir, but not saquinavir at therapeutic levels; in 15 patients, rise in bilirubin occurred in 13 and was more marked in those with Gilbert's TATA box variants [0.8 rising to 2.3 mg/dL] than without [0.5 rising to 0.8 mg/dL]). 11606755
Riddle TM, Kuhel DG, Woollett LA, Fichtenbaum CJ, Hui DY. HIV protease inhibitor induces fatty acid and sterol biosynthesis in liver and adipose tissues due to the accumulation of activated sterol regulatory element-binding proteins in the nucleus. J Biol Chem 2001; 276: 37514-9. (In mice, ritonavir results in increase in plasma triglyceride and cholesterol levels via increase in hydrolysis of precursor sterol regulatory element-binding protein, which causes its release from endoplasmic reticulum and translocation to the nucleus where it induces lipid metabolism enzymes). 11546771
Hill JB, Sheffield JS, Zeeman GG, Wendel GD Jr. Hepatotoxicity with antiretroviral treatment of pregnant women. Obstet Gynecol 2001; 98: 909-11. (Two cases, 28 year old woman on zidovudine, lamivudine and efavirenz developed jaundice at 18 weeks gestation [bilirubin 20.3 mg/dL, ALT 421 U/L], remaining jaundiced until delivered at 27 weeks, resolving in 5 months after delivery; 22 year old started on lamivudine, zidovudine and nelfinavir at 14 weeks gestation and developed jaundice 10 weeks later [bilirubin 8.9 mg/dL, ALT 1598 U/L], progressing to acute liver failure and death). 11704198
Trapé M, Barnosky S. Nelfinavir in expanded postexposure prophylaxis causing acute hepatitis with cholestatic features: two case reports. Infect Control Hosp Epidemiol 2001; 22: 2-3. (Among 15 subjects treated prophylactically with zidovudine, lamivudine and nelfinavir after accidental exposure to HIV, 2 developed symptomatic liver disease; 54 year old physician developed fatigue, nausea, fever and abdominal pain 15 days after starting therapy; 32 year old surgical resident developed fever and nausea at 15 and jaundice after 17 days of therapy. Both resolved within weeks of stopping nelfinavir, continuing others [no laboratory results given]). 11519908
Núñez M, Lana R, Mendoza JL, Martin-Carbonero L, Soriano V. Risk factors for severe hepatic injury after introduction of highly active antiretroviral therapy. J AIDS 2001; 27: 426-31. (Retrospective review of 222 patients started on highly active antiretroviral therapy, 96 with protease inhibitors; 10% had ALT elevations >5 times ULN, risk factors were HCV infection, alcohol use and older age, but not type of agent; transient in all except HCV infected). 11511818
Hernandez LV, Gilson I, Jacobson J, Affi A, Puetz TR, Dindzans VJ. Antiretroviral hepatotoxicity in human immunodeficiency virus-infected patients. Aliment Pharmacol Ther 2001; 15: 1627-32. (Retrospective analysis identified 24 of 65 patients on antiretroviral therapy with suspected hepatotoxicity [ALT twice normal 5 to 90 days after starting or rapid ALT decline with stopping]; risk factors were hepatitis C, older age and low CD4 counts, but not any specific agent or duration of therapy). 11564003
Manegold C, Hannoun C, Wywiol A, Dietrich M, Polywka S, Chiwakata CB, Gunther S. Reactivation of hepatitis B virus replication accompanied by acute hepatitis in patients receiving highly active antiretroviral therapy. Clin Infect Dis 2001; 32: 144-8. (Two cases of reactivation with reappearance of HBsAg in HIV-positive patients with subsequent flare of hepatitis B on antiretroviral therapy; 65 year old man with anti-HBs and anti-HBc without HBsAg, developed HBsAg 4 months after starting antiretroviral therapy [without lamivudine], with transient increase in HBV DNA and ALT followed by resolution; 35 year old man with flare of hepatitis B after withdrawal of lamivudine and subsequent recovery). 11118394
Bonfanti P, Landonio S, Ricci E, Martinelli C, Fortuna P, Faggion I, Quirino T, CISAI Study Group. Risk factors for hepatotoxicity in patients treated with highly active antiretroviral therapy. J Acquir Immune Defic Syndr 2001; 27: 316-8. (Analysis of 1477 Italian patients with HIV infection starting therapy with at least one protease inhibitor; ALT elevations occurred in 5.8 per 100 patient years; ALT levels above 5 times ULN in 2.7 per 100 patient years; risk factors were HCV coinfection and preexisting ALT elevations). 11464155
Monforte AD, Bugarini R, Pezzotti P, De Luca A, Antionori A, Mussini C, Vigevani GM, et al., ICONA Study Group. Low frequency of severe hepatotoxicity and association with HCV coinfection in HIV-positive patients treated with HAART. J Acquir Immune Defic Syndr 2001; 28: 114-23. (Among 1255 patients with HIV infection starting antiretroviral therapy, mean ALT levels did not change and only 4.5% developed ALT above 200 U/L during median follow up of 18 months; the only independent risk factor for ALT elevations was baseline ALT levels). 11588504
Bica I, McGovern B, Char R, Stone D, McGowan K, Scheib R, Snydman DR. Increasing mortality due to end-stage liver disease in patients with HIV infection. Clin Infect Dis 2001; 32: 492-7. (While the mortality rate of HIV infection fell with development of effective antiretroviral therapies, the proportion of deaths due to liver disease has increased from 11.5% in 1991 to 50% in 1999, mostly due to hepatitis C). 11170959
Reisler K. High hepatotoxicity rate seen among HAART patients. AIDS Alert 2001; 16: 118-9. (News report on abstract: study of 10,011 patients in 21 clinical trials with HIV infection, showing that ALT elevations >5 times normal occur in 6.2% of highly active antiretroviral therapy treated patients; 10.8% with efavirenz, 8.9% with nevirapine and 3.6% with delavirdine in short term studies). 11547496
Clark S, Creighton S, Portmann B, Taylor C, Wendon J, Cramp M. Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol 2002; 36: 295-301. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], or nelfinavir, delaviridine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 had signs of hypersensitivity, two had hepatitis B; 5 died, autopsies showing massive necrosis, one with massive steatosis; likely multiple causes). 11830344
Cooper CL, Parbhakar MA, Angel JB. Hepatotoxicity associated with antiretroviral therapy containing dual versus single protease inhibitors in individuals coinfected with hepatitis C virus and human immunodeficiency virus. Clin Infect Dis 2002; 34: 1259-63. (Retrospective analysis of 66 HIV-HCV coinfected patients initiating antiretroviral therapy with protease inhibitors; ALT elevations >5 times ULN occurred in 24% of ritonavir containing vs 22% of ritonavir sparing regimens). 11941553
Stone SF, Lee S, Keane NM, Price P, French MA. Association of increased hepatitis C virus (HCV)-specific IgG and soluble CD26 dipeptidyl peptidase IV enzyme activity with hepatotoxicity after highly active antiretroviral therapy in human immunodeficiency virus-HCV-coinfected patients. J Infect Dis 2002; 186: 1498-502. (Serial testing for levels of anti-HCV [core specific, IgG] and DPP IV enzyme activity in 16 patients with HIV-HCV coinfection on antiretroviral therapy found rises in these markers occurred concurrent with or shortly after ALT elevations thought be suggestive of role of immune reconstitution). 12404169
Dybul M, Fauci AS, Bartlett JG, Kaplan JE, Pau AK; Panel on Clinical Practices for the Treatment of HIV. Guidelines for using antiretroviral agents among HIV-infected adults and adolescents. Recommendations of the Panel on Clinical Practices for Treatment of HIV. MMWR Recomm Rep 2002; 51 (RR-7): 1-55. (Recommendations on use of antiretroviral agents for HIV infection including indications, efficacy, need for monitoring and side effects including hepatotoxicity). 12027060
Chung R, Evans S, Yang Y, Theodore D, Valdez H, Clark R, Shikuma C, et al., AIDS Clinical Trial Group 383 Study Team. Immune recovery is associated with persistent rise in hepatitis C virus RNA, infrequent liver test flares, and is not impaired by hepatitis C virus in co-infected subjects. AIDS 2002; 16: 1915-23. (Analysis of 60 patients with HIV-HCV coinfection starting highly active antiretroviral therapy, HCV RNA levels increased by ~0.4 log IU/mL which persisted to week 48, ALT levels rose early and then fell to baseline, only 2 patients had ALT elevations >5 times ULN, no decompensation). 12351951
Thio CL, Seaberg EC, Skolasky R Jr, Phair J, Visscher B, Muñoz A, Thomas DL; Multicenter AIDS Cohort Study. HIV-1, hepatitis B virus, and risk of liver-related mortality in the Multicenter Cohort Study (MACS). Lancet 2002; 360: 1921-6. (Risk of liver related death was increased in patients with HIV infection and particularly high in those with HIV-HBV coinfection). 12493258
Lemberg DA, Palasanthiran P, Goode M, Ziegler JB. Tolerabilities of antiretrovirals in paediatric HIV infection. Drug Saf 2002; 25: 973-91. (Review of adverse events in children for each of the antiretrovirals; rates of hepatotoxicity appear to be similar in children as adults, mitochondrial toxicity is rare, but deaths due to pancreatitis and liver failure have been reported in children on didanosine). 12408730
Martín-Carbonero L, Núñez M, Ríos P, Pérez-Olmeda M, González-Lahoz J, Soriano V. Liver injury after beginning antiretroviral therapy in HIV/hepatitis C virus co-infected patients is not related to immune reconstitution. AIDS 2002; 16: 1423-5. (Analysis of changes in ALT, CD4 counts, HIV RNA and HCV RNA in 42 HIV/HCV coinfected patients started on antiretroviral therapy; 72% developed ALT elevations, 14% >5 times ULN, but no correlation between amount of HIV decrease or CD4 increase and frequency of ALT elevation, but those with severe injury all had improvements in CD4 counts and slight increase in HCV RNA levels). 12131221
Murcia JM, Boix V, Merino E, Manso MI, Portilla J. Drug toxicity or syndrome of immune restoration causing fulminant cirrhosis after HAART-induced immune recovery. Eur J Clin Microbiol Infect Dis 2002; 21: 153-5. (25 year old man with HIV-HCV-HBV coinfections developed rising ALT levels 1 year after starting stavudine, nelfinavir and nevirapine [peak bilirubin 17.6 mg/dL, ALT 1502 U/L, HCV RNA 786,000 copies/mL, no detectable HBV DNA on several determinations] and acute-on-chronic hepatitis by liver biopsy which progressed to liver failure, despite stopping antivirals and fall of HCV RNA to undetectable; authors attributed acute severe flare to immune reconstitution). 11939401
Shahmanesh M, Cartledge J, Miller R. Lactic acidosis and abnormal liver function in advanced HIV disease. Sex Transm Infect 2002; 78: 139-42. (Case report and discussion: 48 year old man with HIV infection on zidovudine, didanosine and indinavir developed ascites, mild lactemia and abnormal liver tests [ALT 116 U/L, Alk P 324 U/L] and subsequent variceal hemorrhage, multiorgan failure and death, possibly nodular regenerative hyperplasia and not nucleoside analogue related hepatotoxicity). 12081178
Selik R, Byers R, Dworkin M. Trends in diseases reported on US death certificates that mentioned HIV infection. 1987-99. J Acquir Immune Defic Syndr 2002; 29: 378-87. (Analysis of US vital statistics; deaths from AIDS rose from 15,331 in 1987 to 47,977 in 1995 then falling to 16,061 in 1999, with increases in the proportion of deaths due to liver disease from 4.9% in 1987 to 11.6% in 1999). 11917243
Aceti A, Pasquazzi C, Zechini B, De Bac C, LIVERHAART Group. Hepatotoxicity development during antiretroviral therapy containing protease inhibitors in patients with HIV. The role of hepatitis B and C virus infection. J Acquir Immune Defic Syndr 2002; 29: 41-8. (Among 1325 patients starting highly active antiretroviral therapy, 11% developed ALT elevations, 3.2% >5 times ULN, often remaining high at 12 and 24 months; elevations were more common with ritonavir [17.5%], saquinavir [12.6%], and indinavir [8.5%]). 11782588
Núñez M, Rios P, Martin-Carbonero L, Perez-Olmeda M, González-Lahoz J, Soriano V. Role of hepatitis C virus genotype in the development of severe transaminase elevation after the introduction of antiretroviral therapy. J Acquir Immune Defic Syndr 2002; 30: 65-8. (Among 70 patients with HIV-HCV coinfection, 37 [53%] developed ALT elevations after starting antiretroviral therapy, 12 [17%] >5 times ULN, and higher rate in patients with HCV genotype 3 [71% for any elevation; 33% for >5 times ULN]). 12048364
Spengler U, Lichterfeld M, Rockstroh JK. Antiretroviral drug toxicity-a challenge for the hepatologist? J Hepatol 2002; 36: 283-94. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents, with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions). 11830343
Wit FW, Weverling GJ, Weel J, Jurriaans S, Lange JM. Incidence of and risk factors for severe hepatotoxicity associated with antiretroviral combination therapy. J Infect Dis 2002; 186: 23-31. (Retrospective analysis found 6.3% incidence of liver enzyme elevations >5 times ULN among 560 Dutch patients on highly active antiretroviral therapy; 71% had either HBV or HCV infection; risk factors included recent introduction of nevirapine or high dose ritonavir or stopping lamivudine). 12089658
Qurishi N, Kreuzberg C, Luchters G, Effenberger W, Kupfer B, Sauerbruch T, Rockstroh JK, et al. Effect of antiretroviral therapy on liver-related mortality in patients with HIV and hepatitis C virus coinfections. Lancet 2003; 362: 1708-13. (Analysis of liver related mortality in cohort of largely hemophilic patients with HIV infection; 0.45/100,000 in those on highly active antiretroviral therapy vs 0.69 in those on nucleoside analogues only vs 1.70 among antiretroviral untreated patients). 14643119
Carter M. ART and liver-related mortality in HIV/HCV. IAPAC Mon 2003; 9: 315. (News report on the rising proportion of deaths due to liver disease among HIV-infected persons as reported by Qurishi [2003]). 15055165
Dore G. Antiretroviral therapy-related hepatotoxicity: predictors and clinical management. J HIV Ther 2003; 8: 96-100. (Review with suggested algorithm for management of ALT elevations on HAART therapy). 14671507
Weissbrich B, Langmann P, Schubert J, Jassoy C, Klinker H. Resolution of HCV infection in a HIV-infected patient under HAART after several hepatitis flare-ups. Eur J Med Res 2003; 8: 495-8. (Patient with HIV and severe hepatitis C became HCV RNA negative after complications of cirrhosis on long term nevirapine and indinavir therapy). 14644704
Kontorinis N, Dieterich D. Hepatotoxicity of antiretroviral therapy. AIDS Rev 2003; 5: 36-43. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5, grade 2=2.6-5, grade 3=5.1-10, and grade 4=>10 times ULN or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity). 12875106
Lichterfeld M, Fischer HP, Spengler U, Rockstroh JK. [Fatty liver and increased serum lactate in a woman with HIV] Dtsch Med Wochenschr 2003; 128: 81-4. (50 year old developed abdominal pain and hepatomegaly 7 months after starting stavudine, lamivudine, indinavir and low dose ritonavir [ALT 434 U/L, GGT 58 U/L, lactate 9.2 mmol/L, pH 7.2]; liver biopsy showed micro- and macro-steatosis, resolving a few weeks after stopping antivirals; most likely due to stavudine). 12529837
Law WP, Dore GJ, Duncombe CJ, Mahanontharit A, Boyd MA, Ruxrungtham K, Lange JM, et al. Risk of severe hepatotoxicity associated with antiretroviral therapy in the HIV-NAT Cohort, Thailand, 1996-2001. AIDS 2003; 17: 2191-9. (Among 692 patients in 8 controlled trials in Thailand, rate of ALT elevations >5 times ULN was 6.1/100 patient years overall; in multivariate analysis, risk factors were HBV [RR=3.9], HCV [3.0], and use of nonnucleoside reverse transcriptase inhibitors [6.8], rate with nevirapine [18.6/100 person years] higher than efavirenz [2.4]). 14523276
Ofotokun I, Pomeroy C. Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med 2003; 11: 55-9. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men). 12717043
Ogedegbe AO, Sulkowski MS. Antiretroviral-associated liver injury. Clin Liver Dis 2003; 7: 475-99. (Review of hepatotoxicity of antiretrovirals; ALT elevations >5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine, and 8% efavirenz; recommend monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated). 12879995
Livry C, Binquet C, Sgro C, Froidure M, Duong M, Buisson M, Grappin M, et al. Acute liver enzyme elevations in HIV-1-infected patients. HIV Clin Trials 2003; 4: 400-10. (Retrospective analysis of 239 patients with HIV on antiretroviral therapy found ALT or Alk P elevations >2.5 times ULN in 10.7 per 100 patient years in treated and 7.4 per 100 patient years in untreated patients; associated with HCV or HBV co infection, antiretroviral therapy and AIDS severity, but not specific agents). 14628283
Pialoux G, Bonnard P, Rozenbaum W. [Liver toxicity of antiretroviral treatments] Gastroenterol Clin Biol 2003; 27: 155-8. French. (Review of hepatotoxicity of antiretrovirals; elevations in ALT or AST levels above 5 times ULN occur in 5.7% to 18% of patients on combination antiviral therapies). 12658125
Sulkowski MS. Hepatotoxicity associated with antiretroviral therapy containing HIV-1 protease inhibitors. Semin Liver Dis 2003; 23: 183-94. (All 6 protease inhibitors used for HIV infection have been associated with hepatotoxicity, all are extensively metabolized by the hepatic CYP450 system; overall range of ALT elevations above 5 times ULN is 3% to 18%, but symptomatic liver injury occurs in only 1.5 to 5% of patients; risk factors ALT elevations are HCV, HBV and full dose ritonavir). 12800071
Puoti M, Torti C, Ripamonti D, Castelli F, Zaltron S, Zanini B, Spinetti A, et al.; HIV-HCV Co-Infection Study Group. Severe hepatotoxicity during combination antiretroviral treatment: incidence, liver histology, and outcome. J Acquir Immune Defic Syndr 2003; 32; 259-67. (Among 755 HIV-positive patients starting antiretroviral therapy, 26 [4.2/100 person-years] developed ALT elevations above 10 times ULN, but only in patients with HCV [n=25], HBV [n=4] or HDV [n=4] coinfection; 7 died). 12626885
Vennarecci G, Ettorre GM, Antonini M, Maritti M, Moricca P, D'Offizzi G, Narciso P, et al. [Acute liver toxicity of antiretroviral therapy(HAART) after liver transplantation in a patient with HIV-HCV coinfection and associated hepatocarcinoma (HCC)]. Tumori 2003; 89 (4 Suppl): 159-61. Italian. (46 year old man with HIV-HCV coinfection and hepatocellular carcinoma developed severe graft dysfunction immediately after transplant, possibly related to alteration in antiretroviral drug levels). 12903579
Zell SC. Clinical vignette in antiretroviral therapy: jaundice. J Int Assoc Physicians AIDS Care (Chic Ill) 2003; 2: 133-9. (35 year old man with AIDS developed jaundice 17 months after starting lopinavir, stavudine and lamivudine [bilirubin 12.5 mg/dL, ALT 200 U/L, Alk P 435 rising to 958 U/L], resolving in 2 months after substituting nelfinavir for lopinavir). 14986514
Uberti-Foppa C, De Bona A, Morsica G, Galli L, Gallotta G, Boeri E, Lazzarin A. Pretreatment of chronic active hepatitis C in patients coinfected with HIV and hepatitis C virus reduces the hepatotoxicity associated with subsequent antiretroviral therapy. J Acquir Immune Defic Syndr 2003; 33: 146-52. (Rates of ALT elevations >5 times ULN or 3.5 times baseline were less among 66 patients who were pretreated for hepatitis C [interferon with or without ribavirin] compared to 39 who were not treated [6% vs 15%, p=NS]). 12794546
French AL, Benning L, Anastos K, Augenbraun M, Nowicki M, Sathasivam K, Terrault NA. Longitudinal effect of antiretroviral therapy on markers of hepatic toxicity: impact of hepatitis C coinfection. Clin Infect Dis 2004; 39: 402-10. (Statistical analysis of ALT and AST levels in 1106 HIV infected women who initiated highly active antiretroviral therapy; proportion with elevations was higher in HIV coinfected, but did not increase in either group or by agent class used after starting therapy). 15307009
Sulkowski MS, Mehta SH, Chaisson RE, Thomas DL, Moore RD. Hepatotoxicity associated with protease inhibitor-based antiretroviral regimens with or without concurrent ritonavir. AIDS. 2004; 18: 2277-84. (Prospective analysis of 1161 patients [1996-2003] started on protease inhibitors, ALT >5 times ULN occurred in 12.7%, with slightly higher rates for saquinavir/ritonavir [17.2%] and with HCV coinfection; multivariate analysis identified HCV infection and use of saquinavir or indinavir associated with ALT >5 times ULN). 15577540
Meraviglia P, Schiavini M, Castagna A, Viganò P, Bini T, Landonio S, Danise A, et al. Lopinavir/ritonavir treatment in HIV antiretroviral-experienced patients: evaluation of risk factors for liver enzyme elevation. HIV Med 2004; 5: 334-43. (Among 782 HIV-positive patients treated with lopinavir and low dose ritonavir, 71 [9%] developed abnormal liver tests, mostly mild, asymptomatic and self-limited, but 4 had symptomatic hepatitis, 3 were jaundiced and one died; multivariate analysis showed HCV and HBV coinfection, younger age, high ALT values and use of efavirenz were risk factors for abnormal liver tests). 15369508
Gathe JC Jr, Ive P, Wood R, Schümann D, Bellos NC, DeJesus E, Gladysz A, et al. SOLO: 48-week efficacy and safety comparison of once-daily fosamprenavir /ritonavir versus twice-daily nelfinavir in naive HIV-1-infected patients. AIDS 2004; 18: 1529-37. (In a controlled trial of fosamprenavir with low dose ritonavir versus nelfinavir, both combined with abacavir and lamivudine, ALT elevations above 5 times ULN occurred in 8% of both treatment arms). 15238771
Eholié SP, Lacombe K, Serfaty L, Wendum D, Girard PM. Acute hepatic cytolysis in an HIV-infected patient taking atazanavir. AIDS 2004; 18: 1610-1. (56 year old woman developed fatigue and ALT elevations 7 months after being switched from lopavir/r and stavudine to atazanavir and tenofovir while remaining on didanosine [bilirubin normal, ALT 405 U/L, Alk P 158 U/L], resolving 8 weeks after stopping atazanavir, subsequently tolerating didanosine, tenofovir and nelfinavir). 15238786
González de Requena D, Núñez M, Jiménez-Nácher I, González-Lahoz J, Soriano V. Liver toxicity of lopinavir-containing regimens in HIV-infected patients with or without hepatitis C coinfection. AIDS Res Hum Retroviruses 2004; 20: 698-700. (Among 120 patients started on lopinavir-containing regimens for HIV, ALT elevations above 5 times ULN or above 3.5 times baseline arose in 6 [5%], all cases occurring in HCV infected [n=4] or patients abusing alcohol [n=2]). 15307912
Kottilil S, Polis MA, Kovacs JA. HIV Infection, hepatitis C infection, and HAART: hard clinical choices. JAMA 2004; 292: 243-50. (Case report of patient with HIV and HCV coinfection on antiretrovirals; nonresponse to a course of peginterferon and ribavirin). 15249574
Hicks C, King MS, Gulick R, Clinton White A, Eron JJ, Kessler HA, Benson C, et al. Long-term safety and durable antiretroviral activity of lopinavir/ritonavir in treatment-naï patients: 4-year follow up study. AIDS 2004; 18: 775-9. (Among 100 treatment-naïve patients treated with lopinavir with low dose ritonavir in differing doses, ALT elevations >5 times ULN occurred in 11% by 4 years; rates were higher in those with HBV or HCV coinfection). 15075512
Sulkowski MS. Drug-induced liver injury associated with antiretroviral therapy that includes HIV-1 protease inhibitors. Clin Infect Dis 2004; 38 Suppl 2: S90-7. (Review focusing upon protease inhibitors; forms of injury include indirect hyperbilirubinema caused by indinavir and atazanavir and ALT elevations that occur in 3% to 11% of patients treated with combinations including protease inhibitors, higher rates of ALT elevations are associated with HBV and HCV coinfection, full dose ritonavir, alcohol abuse and during initial therapy accompanied by marked rises in CD4 counts). 14986280
Te HS. Cholestasis in HIV-infected patients. Clin Liver Dis 2004; 8: 213-28, viii-ix. (Review of causes of cholestasis in HIV infected patients including antiretrovirals). 15062202
Havlir DV, O'Marro SD. Atazanavir: new option for treatment of HIV infection. Clin Infect Dis 2004; 38: 1599-1604. (Atazanavir was the 7th protease inhibitor approved for use and given with ritonavir boost [300/100 mg] once daily, metabolized by and inhibits CYP 3A and UGT1A1, bilirubin levels >2.6 times ULN occur in 1/3 of patients, ALT elevations >5 times ULN in 9% to 15% of patients with HBV or HCV co-infection, rates of enzyme elevations were similar to comparative agents). 15156449
Verucchi G, Calza L, Biagetti C, Attard L, Costigliola P, Manfredi R, Pasquinelli G, et al. Ultrastructural liver mitochondrial abnormalities in HIV/HCV-coinfected patients receiving antiretroviral therapy. J Acquir Immune Defic Syndr 2004; 35: 326-8. (Electron microscopy of 34 liver biopsies done on HIV-HCV coinfected patients on long term antiretroviral therapy [2-14 years] and in 4 on no therapy found mitochondrial abnormalities in all except 1, but not associated with a specific antiviral agent and unclear whether due to therapy, HCV, HIV or other factors). 15076252
Sherman KE, Shire NJ, Cernohous P, Rouster SD, Omachi JH, Brun S, Da Silva B. Liver injury and changes in hepatitis C Virus (HCV) RNA load associated with protease inhibitor-based antiretroviral therapy for treatment-naive HCV-HIV-coinfected patients: lopinavir-ritonavir versus nelfinavir. Clin Infect Dis 2005; 41: 1186-95. (Among 70 patients with HIV-HCV coinfection treated with lopinavir/ritonavir [r] vs nelfinavir for 48 weeks, slight increase in HCV RNA levels, particularly in those with low initial CD4 counts occurred and were associated with ALT flares above 5 times ULN in 19.5% of nelfinavir vs 7% of lopinavir/r treated patients). 16163639
Abrescia N, D'Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. Hepatotoxicity of antiretroviral drugs. Curr Pharm Des 2005; 11: 3697-710. (Review of hepatotoxicity of antiretrovirals; recommended approach to managing patients with elevations in ALT levels during therapy). 16305505
Anon. Drug-induced hepatitis with saquinavir/ritonavir + rifampin. AIDS Clin Care 2005; 17: 32. (News report that Roche sent an alert letter reporting that 11 of 28 healthy controls developed ALT elevations in a phase 1 study of saquinavir/ ritonavir with rifampin [Schmitt, 2009]). 15828118
Kramer J, Giordano T, Soucheck J, El-Serag H. Hepatitis C coinfection increases the risk of fulminant hepatic failure in patients with HIV in the HAART era. J Hepatol 2005; 42: 309-14. (Analysis of US Veterans Administration hospital database, including 16,439 HIV-positive patients, identified 92 patients with acute liver failure [0.5 per 1000 patient-years], risk factors were HCV coinfection, but casees occurred only during the highly active antiretroviral therapy era). 15710213
Salmon-Ceron D, Lewden C, Morlat P, Bevilacqua S, Jougla E, Bonnet F, Heripret L, et al., the Morality 2000 Study Group. Liver disease as a major cause of death among HIV infected patients; role of hepatitis C and B viruses and alcohol. J Hepatol 2005; 42: 799-805. (In analysis of 924 deaths during 2000 among HIV infected patients in France; liver disease accounted for 11% of all deathsl, 31% among HCV coinfected, 20% HBV coinfected, but only 2% in patients without HBV or HCV; 88% of liver deaths were from end stage liver disease and 15% had hepatocellular carcinoma; the authors estimated that only 9% of liver disease deaths were attributable to drug hepatotoxicity). 15973779
Bonfanti P, Ricci E, Penco G, Orofino G, Bini T, Sfara C, Miccolis S, et al., CISAI Study Group. Low incidence of hepatotoxicity in a cohort of HIV patients treated with lopinavir/ritonavir. AIDS 2005; 19: 1433-4. (Among 755 patients with HIV receiving lopinavir/ritonavir followed in an Italian surveillance program, 0.59% per year had ALT elevations >5 times ULN, a lower rate than in most studies). 16103779
Mocroft A, Soriano V, Rockstroh J, Reiss P, Kirk O, de Wit S, Gatell J, et al.; EuroSIDA Study Group. Is there evidence for an increase in the death rate from liver-related disease in patients with HIV? AIDS 2005; 19: 2117-25. (Among ~11,000 patients followed in European studies of HIV infected subjects, 184 [1.7%] had liver related death, decreasing by 7% between 1995 and 2004; controlling for CD4 count and patient characteristics [but not age or duration of infection], however, liver related death rate has increased). 16284461
Mehta SH, Thomas DL, Torbenson M, Brinkley S, Mirel L, Chaisson RE, Moore RD, et al. The effect of antiretroviral therapy on liver disease among adults with HIV and hepatitis C coinfection. Hepatology 2005; 41: 123-31. (Analysis of liver biopsy histology from 210 patients with HIV-HCV coinfection; neither fibrosis nor necroinflammatory activity correlated with episodes of liver enzyme elevations due to antiretroviral therapy; predictors of fibrosis included persistent ALT elevations, age and alcohol use). 15619237
Núñez M, Soriano V. Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. Drug Saf 2005; 28: 53-66. (Review of liver toxicity of antiretrovirals). 15649105
Flexner C, Bate G, Kirkpatrick P. Tipranavir. Nat Rev Drug Discov 2005; 4: 955-6. (Review of discovery, structure, activity, clinical efficacy, indications and "market analysis" of tipranavir). 16370086
Aranzabal L, Casado JL, Moya J, Quereda C, Diz S, Moreno A, Moreno L, et al. Influence of liver fibrosis on highly active antiretroviral therapy-associated hepatotoxicity in patients with HIV and hepatitis C virus coinfection. Clin Infect Dis 2005; 40: 588-93. (Among 107 patients with HIV-HCV coinfection with liver histology, 27 [25%: 5 events per 100 patient years] had ALT elevations >5 times ULN or >3.5 times baseline; more frequent in patients with higher levels of fibrosis [38% vs 15%], also higher in patients receiving nonnucleoside reverse transcriptase inhibitors). 15712082
Servin-Abad L, Molina E, Baracco G, Arosemena L, Regev A, Jeffers L, Schiff E. Liver enzyme elevation after HAART in HIV-HCV co-infection. J Viral Hepat 2005; 12: 429-34. (Among 85 patients with HIV-HCV coinfection who started antiretroviral therapy and were followed for at least 1 year, 4% per year developed ALT or AST elevations >5 times ULN, more frequent with higher baseline levels; all asymptomatic and no association with a specific agent). 15985015
Torti C, Lapadula G, Casari S, Puoti M, Nelson M, Quiros-Roldan E, Bella D, et al.; EPOKA-MASTER Study Group. Incidence and risk factors for liver enzyme elevation during highly active antiretroviral therapy in HIV-HCV co-infected patients: results from the Italian EPOKA-MASTER Cohort. BMC Infect Dis 2005; 5: 58. (Among 1038 HIV-HCV coinfected patients starting antiretroviral therapy, risk of ALT elevations >5 times ULN was 17.1 per 100 patient years in treatment-naïve and 8.2 in treatment-experienced patients; risk factors for elevations were baseline ALT levels and nonnucleoside reverse transcriptase inhibitor use). 16018804
Rotger M, Taffe P, Bleiber G, Gunthard HF, Furrer H, Vernazza P, Drechsler H, et al.; Swiss HIV Cohort Study. Gilbert syndrome and the development of antiretroviral therapy-associated hyperbilirubinemia. J Infect Dis 2005; 192: 1381-6. (Retrospective analysis of 96 Swiss patients with HIV infection genotyped for UGT1A1 and assessed for bilirubin elevations during antiretroviral therapy; total bilirubin increased by 0.43 on atazanavir and 0.28 on indinavir, and higher levels with hetero- or homo-zygosity for UGT1A1 *28). 16170755
Sulkowski MS, Mehta SH, Torbenson M, Afdhal NH, Mirel L, Moore RD, Thomas DL. Hepatic steatosis and antiretroviral drug use among adults coinfected with HIV and hepatitis C virus. AIDS 2005; 19: 585-92. (Analysis of liver histology from 112 patients with HIV-HCV coinfection; 40% had some degree of steatosis, which was independently associated with white race, body weight, high blood sugar and ever having used stavudine). 15802977
Verma S, Bhakta H, Nowain A, Pais S, Kanel G, Squires K, Squires K. Severe cholestatic liver injury days after initiating antiretroviral therapy in a patient with AIDS: drug toxicity or immune reconstitution inflammatory syndrome? Dig Dis Sci 2005; 50: 1813-7. (37 year old man with AIDS developed rash and fever one week after starting efavirenz and lopinavir/ritonavir and one day after restarting azithromycin, trimethoprim/sulfamethoxazole [TMP/SMS], one week later became jaundiced [bilirubin 0.4 rising to 9.9 mg/dL, ALT 103 U/L and Alk P 700 U/L], values normalizing in a few weeks, and jaundice recurring after 2 rechallenges using same antiretroviral regimen without TMP/SMS). 16187179
Canta F, Marrone R, Bonora S, D'Avolio A, Sciandra M, Sinicco A, De Rosa FG, et al. Pharmacokinetics and hepatotoxicity of lopinavir/ritonavir in non-cirrhotic HIV and hepatitis C virus (HCV) co-infected patients. J Antimicrob Chemother 2005; 55: 280-1. (Among 149 HIV infected patients started on lopinavir with low dose ritonavir, 78 were HCV coinfected and cumulative rates of ALT elevations above 2 times ULN were 12.5% in monoinfected vs 61% in coinfected patients and degree of elevations were lower in those without HCV infection; those with and without ALT elevations had similar peak drug levels). 15650005
Aceti A, Pasquazzi C, Zechini B, De Bac C; the LIVERHAART Group. Development of hepatotoxicity in HIV patients switching at least one protease inhibitor. Int J STD AIDS 2005; 16: 148-52. (Among 182 patients with HIV infection on at least one protease inhibitor for at least 24 months and who then switched to another agent, ALT levels above 5 times ULN occurred in 40% on ritonavir, 18% nelfinavir, 12% indinavir, 11% saquinavir; thus, switching protease inhibitors was not always followed by similar ALT increases on new agent). 15825250
Rabaud C, Burty C, Grandidier M, Christian B, Penalba C, Béinot I, Jeanmaire H, et al. Tolerability of postexposure prophylaxis with the combination of zidovudine-lamivudine and lopinavir-ritonavir for HIV infection. Clin Infect Dis 2005; 40: 303-5. (Among 121 persons given zidovudine, lamivudine, lopinavir/ritonavir for prevention of HIV after acute exposure, nausea occurred in 67%, fatigue 47%, rash 11%, ALT elevations >3 times ULN in 4%). 15655751
Bruno R, Sacchi P, Maiocchi L, Zocchetti C, Filice G. Hepatotoxicity and nelfinavir: a meta-analysis. Clin Gastroenterol Hepatol 2005; 3: 482-8. (Pooled analysis of 4268 patients in 4 clinical trials, combined estimates of liver related enzyme level increases were 2.9% for nelfinavir, 3.1% indinavir, 5.4% saquinavir, 9.6% ritonavir, and 12% for saquinavir/r based regimens). 15880318
Mira JA, Macias J, Giron-Gonzalez JA, Merino D, Gonzales-Serrano M, Jimenez-Mejias ME, Caballero-Granado FJ, et al. Incidence of and risk factors for severe hepatotoxicity of nelfinavir-containing regimens among HIV-infected patients with chronic hepatitis C. J Antimicrob Chemother 2006; 58: 140-6. (Among 80 patients with HIV-HCV coinfection treated with nelfinavir, 9 had an episode of hepatotoxicity, 8 with ALT levels above 5 times ULN and one had hepatic decompensation; nevirapine use was associated with a higher risk of hepatic side effects [8.9]). 16720565
Manfredi R, Sabbatani S. Serious, multi-organ hypersensitivity to lopinavir alone, involving cutaneous-mucous rash, and myeloid, liver, and kidney function. AIDS 2006; 20: 2399-400. (38 year old woman developed Stevens Johnson syndrome 5 days after reintroduction of antiretroviral therapy using lamivudine, stavudine and lopinavir/ritonavir, lopinavir being the only new agent; with pancytopenia, renal dysfunction and increase in liver tests which resolved within 15 days of stopping and did not recur on atazanavir/ritonavir based regimen). 17117031
Julg B, Bogner JR, Goebel FD. Severe hepatotoxicity associated with the combination of enfuvirtide and tipranavir/ritonavir: case report. AIDS 2006; 20: 1563. (52 year old man with HIV-HBV co-infection developed marked increase in ALT [538 U/L] without jaundice, 2 weeks after adding tipranavir and ritonavir to a regimen of zidovudine, lamivudine and enfuvirtide, resolving within 4 weeks of stopping; possibly related to effects of enfuvirtide on drug levels, no analysis of HBV reactivation or lamivudine resistance). 16847416
Pineda JA, Palacios R, Rivero A, Abdel-Kader L, Márquez M, Cano P, Mira JA, et al. Low incidence of severe liver toxicity in patients receiving antiretroviral combinations including atazanavir. J Antimicrob Chemother 2006; 57: 1016-7. (Among 99 patients with HIV started on atazanavir, 3 developed a severe liver event, 2 with decompensation and one with ALT elevations above 5 times ULN, all 3 were either HBV or HCV coinfected). 16556636
Shelton MJ, Wire MB, Lou Y, Adamkiewicz B, Min SS. Pharmacokinetic and safety evaluation of high-dose combinations of fosamprenavir and ritonavir. Antimicrob Agents Chemother 2006; 50: 928-34. (Pharmacokinetic studies of fosamprenavir, a prodrug of amprenavir, combined with low dose ritonavir; increased rates of ALT elevations with higher doses [32% vs 4% and 12% with lower doses in a 14 day trial]). 16495253
Servoss JC, Kitch DW, Andersen JW, Reisler RB, Chung RT, Robbins GK. Predictors of antiretroviral-related hepatotoxicity in the adult AIDS Clinical Trial Group (1989-1999). J Acquir Immune Defic Syndr 2006; 43: 320-3. (In an analysis of factors predicting "serious hepatotoxicity" that arose in 9% of 8851 patients with HIV infection enrolled in trials of antiretroviral therapy, factors identified included baseline liver test abnormalities, HCV infection, and in subgroups, didanosine, nevirapine and stavudine). 16967041
Hofman P, Nelson AM. The pathology induced by highly active antiretroviral therapy against human immunodeficiency virus: an update. Curr Med Chem 2006; 13: 3121-32. (Review of pathology of adverse effects of antiretroviral agents with examples of mitochondrial liver injury and cholestasis). 17168701
Núñez M. Hepatotoxicity of antiretrovirals: incidence, mechanisms and management. J Hepatol 2006; 44 (1 Suppl): S132-9. (Review of hepatotoxicity of antiretrovirals mentions that elevations of ALT or AST levels above 5 times ULN occur in 2-18% of HIV-positive patients starting therapy, elevations being more frequent with HCV or HBV coinfection; combination of protease inhibitors with low dose ritonavir does not seem to increase risk; agents with highest risk are nevirapine and other nonnucleoside reverse transcriptase inhibitors). 16364487
Palacios R, Vergara S, Rivero A, Aguilar I, Mací J, Camacho A, Lozano F, et al. Low incidence of severe liver events in HIV patients with and without hepatitis C or B coinfection receiving lopinavir/ritonavir. HIV Clin Trials 2006; 7: 319-23. (Retrospective analysis of 388 patients with HIV infection starting antiretroviral regimens, that included lopinavir with low dose ritonavir, identified 6 cases of severe liver injury, all in HCV coinfected patients and arising within first 6 months of treatment for a rate of ~1% per year). 17197379
Torti C, Lapadula G, Puoti M, Casari S, Uccelli MC, Cristini G, Bella D, et al. Influence of genotype 3 hepatitis C coinfection on liver enzyme elevation in HIV-1-positive patients after commencement of a new highly active antiretroviral regimen: results from the EPOKA-MASTER Cohort. J Acquir Immune Defic Syndr 2006; 41: 180-5. (Analysis of 492 HIV-HCV coinfected patients treated with highly active antiretroviral therapy found ALT elevations >5 times ULN in 14 per 100 patient years, higher in those with genotype 3 [25] compared to other genotypes [11]; patients with genotype 3 also had higher ALT levels). 16394850
Jain MK, Parekh NK, Hester J, Lee WM. Aminotransferase elevation in HIV/hepatitis B virus co-infected patients treated with two active hepatitis B virus drugs. AIDS Patient Care STDS 2006; 20: 817-22. (3 cases of transient flare of hepatitis B and loss of HBeAg after initiation of tenofovir, lamivudine and protease inhibitor in HIV-HBV coinfected patients with preexisting HBeAg and high levels of HBV DNA; ALT 892, 691 and 328 U/L and bilirubin 3.5, 5.8 and normal; 2 were IgM anti-HBc positive; all resolved on continuing therapy). 17192146
Sauleda S, Martorell M, Esteban JI, Tural C, Ruiz I, Puig L, Esteban R, et al. Hepatotoxicity of antiretroviral drugs in HIV HCV patients with congenital coagulopathies followed at a Haemophilia Unit during a decade. Haemophilia 2006; 12: 228-36. (Retrospective analysis of 246 courses of antiretroviral therapy in 47 patients with hemophilia and HIV infection; ALT elevations >5 times ULN occurred during 28 treatment courses [11%]; most were asymptomatic; one death from liver failure in patient with cirrhosis). 16643206
Hicks CB, Cahn P, Cooper DA, Walmsley SL, Katlama C, Clotet B, Lazzarin A, et al.; RESIST investigator group. Durable efficacy of tipranavir-ritonavir in combination with an optimized background regimen of antiretroviral drugs for treatment-experienced HIV-1-infected patients at 48 weeks in the Randomized Evaluation of Strategic Intervention in multi-drug resistant patients with Tipranavir (RESIST) studies: an analysis of combined data from two randomized open-label trials. Lancet 2006; 368: 466-75. (Trial of tipranavir/ritonavir versus comparator protease inhibitors for 48 weeks in 1483 patients with HIV infection; overall rates of side effects were similar in two arms; rates of ALT elevations >5 times ULN were 10.2% in tipranavir/ritonavir and 3.3% in comparator arms; no mention of clinically apparent liver injury, hepatitis or deaths from liver disease). 16890833
Brau N, Salvatore M, Rios-Bedoya CF, Fernandez-Carbia A, Paronetto F, Rodriguez-Orengo JF, Rodriguez-Torres M. Slower fibrosis progression in HIV/HCV-coinfected patients with successful HIV suppression using antiretroviral therapy. J Hepatol 2006; 44: 47-55. (Comparison of liver histology and estimated fibrosis progression rate among 274 patients with HIV-HCV coinfection vs 382 with HCV infection alone; rate was higher in HIV infected, but only if HIV RNA was detectable). 16182404
Maida I, Babudieri S, Selvia C, D'Offizi G, Fenu L, Solinas G, Narciso P, et al. Liver enzyme elevation in hepatitis C virus (HCV)-HIV-coinfected patients prior to and after initiating HAART: role of HCV genotypes. AIDS Res Hum Retorviruses 2006; 22: 139-143. (Analysis of 306 HIV-positive patients starting antiretroviral therapy [48% with HCV coinfection], only 5 [4%] had ALT elevations above 5 times ULN, all with preexisting ALT elevations; 2 [5.1%] with HCV genotype 3 and 2 [2.3%] with other HCV genotypes). 16478395
Cicconi P, Cozzi-Lepri A, Phillips A, Puoti M, Antonucci G, Manconi PE, Tositti G, et al. for the ICoNA Study Group. Is the increased risk of liver enzyme elevation in patients co-infected with HIV and hepatitis virus greater in those taking antiretroviral therapy? AIDS 2007; 21: 599-606. (Among 5272 patients in an Italian observational study [47% with HCV or HBV coinfection], 275 developed ALT elevations above 5 times ULN or 3.5 times baseline [15 per 1000 person-years], coinfection increased risk of elevations [relative risk: RR=5.1], but not highly active antiretroviral therapy [RR=1.19]). 17314522
Bourlière M, Duclos-Vallée JC, Pol S. [Liver and antiretrovirals: hepatotoxicity, steatosis and monitoring of patients with liver disease] Gastroenterol Clin Biol 2007; 31: 895-905. French. (Review of hepatotoxicity of antiretrovirals discussing patterns of toxic idiosyncrasy, hypersensitivity [nevirapine and abacavir], mitochondrial toxicity [zalcitabine, didanosine, stavudine and zidovudine], steatohepatitis [protease inhibitors with lipodystrophy], immune restoration [in patients with HIV-HBV or -HCV coinfection]; provides recommendations for management focusing on prevention and monitoring). 18166875
Raffi F, Battegay M, Rusconi S, Opravil M, Blick G, Steigbigel RT, Kraft M, et al. Combined tipranavir and enfuvirtide use associated with higher plasma tipranavir concentrations but not with increased hepatotoxicity: sub-analysis from RESIST. AIDS 2007; 21:1 977-80. (Analysis of clinical trial of tipranavir/ritonavir [r] vs comparator protease inhibitors/r who received enfuvirtide; tipranavir [+31%], lopinavir [+19%] and saquinavir levels [39%] were higher in enfuvirtide treated, but rates of ALT elevations above 5 times ULN were lower with each agent [6.5% vs 13%; 1% vs 2.5%; 0.9% vs 1.6%] 17721109
Rachlis A, Clotet B, Baxter J, Murphy R, Lefebvre E. Safety, tolerability, and efficacy of darunavir (TMC114) with low-dose ritonavir in treatment-experienced, hepatitis B or C co-infected patients in POWER 1 and 3. HIV Clin Trials 2007; 8: 213-20. (Pooled analysis of two trials of darunavir with low dose ritonavir in 697 HIV infected patients; rate of ALT elevations similar in darunavir/r treated vs other protease inhibitor treated, any elevation in 23% vs 24% and >5 times ULN in 1.7% vs 2.0% of those without coinfection; higher rates with co-infection 5.1% vs 10%). 17720661
de Mendoza C, Morelló J, Garcia-Gascó P, Rodríguez-Novoa S, Soriano V. Tipranavir: a new protease inhibitor for the treatment of antiretroviral-experienced HIV-infected patients. Expert Opin Pharmacother 2007; 8: 839-50. (Review of tipranavir; a nonpeptidic protease inhibitor, used in salvage therapy always given in combination with low dose ritonavir [r], ALT elevations above 5 times ULN occur in 10% of tipranavir/r vs 3% in comparator protease inhibitor/r treated patients, and rates with tipranavir alone are similar to tipranavir/r; in addition, cases of clinically apparent liver injury and hepatic decompensation have been reported). 17425479
Pavel S, Burty C, Alcaraz I, de la Tribonnière X, Baclet V, Ajana F, Mouton Y, et al. Severe liver toxicity in postexposure prophylaxis for HIV infection with a zidovudine, lamivudine and fosamprenavir/ritonavir regimen. AIDS 2007; 21: 268-9. (Among 26 HIV-negative subjects given prophylaxis against HIV infection after acute exposure using zidovudine, lamivudine and fosamprenavir/ritonavir for 4 weeks, 7 developed abdominal pain and nausea, three had rash and two had ALT increases at week 1 [with rash, ALT 958 U/L] and week 2 [with nausea, ALT 517 U/L], resolving rapidly upon stopping). 17197833
Chauvel O, Lacombe K, Bonnard P, Lascoux-Combe C, Molina J-M, Miailhes P, Girard P-M, et al. Risk factors for acute liver enzyme abnormalities in HIV-hepatitis B virus-coinfected patients on antiretroviral therapy. Antivir Ther 2007; 12: 1115-26. (Analysis of 300 French patients with HIV-HBV coinfection during antiretroviral therapy, rate of ALT or AST elevations above 2 times ULN was 14 per 100 person years; rate of ALT, Alk P and bilirubin elevations above 2 times ULN was 7 per 100 person-years; independent risk factors for ALT elevations were higher HBV DNA and HIV RNA levels and higher CD4 counts, but not specific agents; risk factors for cholestatic injury were duration of HIV infection, protease inhibitor use and recent change in regimen). 18018770
Chihrin S, Antoniou T, Raboud J, Shen S, Govan V, Fletcher D, Rachlis A, et al. Risk factors for grade 3-4 liver enzyme elevation in HIV and hepatitis C coinfected patients on combination antiretroviral therapy. AIDS Patient Care STDS 2007; 21: 469-78. (Retrospective analysis of risk factors for ALT elevations above 5 times ULN in 23% of 151 HIV-HCV coinfected patients starting new antiretroviral regimen identified lopinavir/r as associated with a higher rate of elevations, but baseline aminotransferase values were often not available). 17651028
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. Side effects of HIV therapy. J Dtsch Dermatol Ges 2007; 5: 745-54. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide] and hyperpigmentation [zidovudine, emtricitabine]). 17760894
Gil ACM, Lorenzetti R, Mendes GB, Marcillo AM, Toro AADC, da Silva MTN, dos Santos Vilela MM. Hepatotoxicity in HIV-infected children and adolescents on antiretroviral therapy. Sao Paulo Med J 2007; 125: 205-9. (In a retrospective analysis of 152 children [ages 1 to 18 years] with HIV on antiretroviral therapy, only 14 [10%] had ALT elevations and all were less than 5 times ULN; 4 were also on antituberculosis therapy; rarely used nonnucleoside reverse transcriptase inhibitors). 17992389
Jain MK. Drug-induced liver injury associated with HIV medications. Clin Liver Dis 2007; 11: 615-39, vii-viii. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]). 17723923
Molina JM, Cohen C, Katlama C, Grinsztejn B, Timerman A, Pedro Rde J, Vangeneugden T, et al.; TMC114-C208 study Group; TMC114-C215 Study Group. Safety and efficacy of darunavir(TMC114) with low-dose ritonavir in treatment-experienced patients: 24-week results of POWER 3. J Acquir Immune Defic Syndr 2007; 46: 24-31. (Open labeled study of darunavir/ritonavir [r] in combination with optimized background regimen for 24 weeks in 246 treatment-experienced patients with HIV infection; ALT elevations above 5 times ULN occurred in 8 patients [2%] and there was no clinically apparent hepatotoxicity or deaths from liver disease). 17621237
Madruga JV, Berger D, McMurchie M, Suter F, Banhegyi D, Ruxrungtham K, Norris D, Lefebvre E, et al.; TITAN study group. Efficacy and safety of darunavir-ritonavir compared with that of lopinavir-ritonavir at 48 weeks in treatment-experienced, HIV-infected patients in TITAN: a randomised controlled phase III trial. Lancet 2007; 370: 49-58. (In a trial of darunavir/ritonavir[r] versus lopinavir/r combined with optimized background regimens for 48 weeks in 595 patients with HIV infection, ALT elevations occurred in 9% of both groups; no mention of clinically apparent hepatitis and no liver related deaths). 17617272
Clotet B, Bellos N, Molina JM, Cooper D, Goffard JC, Lazzarin A, Wöhrmann A, et al.; POWER 1 and 2 study groups. Efficacy and safety of darunavir-ritonavir at week 48 in treatment-experienced patients with HIV-1 infection in POWER 1 and 2: a pooled subgroup analysis of data from two randomised trials. Lancet 2007; 369: 1169-78. (Trial of darunavir/ritonavir versus comparator protease inhibitors in antiretroviral regimen for 48 weeks in 230 patients with HIV infection; ALT elevations above 5 times ULN occurred in 2% of darunavir/ritonavir vs 3% of comparator treated patients; no mention of clinically apparent liver injury in list of adverse reactions). 17416261
Labarga P, Soriano V, Vispo ME, Pinilla J, Martin-Carbonero L, Castellares C, Casado R, et al. Hepatotoxicity of antiretroviral drugs is reduced after successful treatment of chronic hepatitis C in HIV-infected patients. J Infect Dis 2007; 196: 670-6. (Among 133 patients with HIV-HCV coinfection who were treated with interferon or peginterferon, 33% had a sustained response and subsequent yearly rate of hepatic events was higher among nonresponders [12.9%] than responders [3.1%]; also more common with receipt of di-deoxynucleosides). 17674307
Mussi-Pinhata MM, Rego MA, Freimanis L, Kakehasi FM, Machado DM, Cardoso EM, Read JS.; NISDI Perinatal Protocol Study Group. Maternal antiretrovirals and hepatic enzyme, hematologic abnormalities among human immunodeficiency virus type 1-uninfected infants: the NISDI perinatal study. Pediatr Infect Dis J 2007; 26: 1032-7. (Analysis of liver enzyme elevations in newborns of HIV infected mothers on various antiretroviral regimens, found that infants whose mothers received protease inhibitors were more likely to have ALT elevations [odds ratio 1.9], similarly for nonnucleoside reverse transcriptase inhibitors [odds ratio 2.4], most elevations were mild and self-limited). 17984811
Rosenthal E, Pialoux G, Bernard N, Pradler C, Rey D, Bentata M, Michelet C, et al.; GERMIVIC Joint Study Group. Liver-related mortality in human-immunodeficiency-virus-infected patients between 1995 and 2003 in the French GERMIVIC Joint Study Group Network (MORTAVIC 2003 Study). J Viral Hepat 2007; 14: 183-8. (A rising proportion of deaths among HIV infected patients in France were due to end stage liver disease: 1.5% in 1995, 6.6% in 1997, 14.3% in 2001 and 12.6% in 2003, HCV being the major cause [93%] and high alcohol intake frequently present [26%]). 17305884
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Recommendations on use of antiviral therapy in adults with HIV infection including use of several agents that had been recently approved: raltegravir, maraviroc and etravirine). 18677028
Bae WH, Wester C, Smeaton LM, Shapiro RL, Lockman S, Onyait K, Thior I, et al. Hematologic and hepatic toxicities associated with antenatal and postnatal exposure to maternal highly active antiretroviral therapy among infants. AIDS 2008; 22: 1633-40. (Among 69 newborns exposed to antiretrovirals in utero, only 1 had ALT elevations above 10 times ULN, compared to 0 of 109 unexposed newborns). 18670224
Inductivo-Yu I, Bonacini M. Highly active antiretroviral therapy-induced liver injury. Current Drug Safety 2008; 3: 4-13. (Review of drug induced liver injury due to antiretroviral agents). 18690975
Jevtovi. DJ, Ranin J, Salemovi. D, Pesic I, Dragovic G, Zerjav S, Djurkovic-Djakovic O. The prevalence and risk of hepatitis flares in a Serbian cohort of HIV and HCV co-infected patients treated with HAART. Biomed Pharmacother 2008; 62: 21-5. (Among 364 HIV infected patients treated with antiretrovirals in Belgrade between 1998-2006, 24 [7%] developed ALT elevations above 5 times ULN [mostly asymptomatic], risk factors for elevations being HCV coinfection [21] and use of stavudine and saquinavir/ritonavir). 17223307
Akhtar MA, Mathieson K, Arey B, Post J, Prevette R, Hillier A, Patel P, et al. Hepatic histopathology and clinical characteristics associated with antiretroviral therapy in HIV patients without viral hepatitis. Eur J Gastroenterol Hepatol 2008; 20: 1194-204. (Among 23 patients with HIV infection without HBV or HCV coinfection who had with abnormal liver tests, 17 [74%] were attributed to antiretroviral agents [defintely in 6, possibly in 11]; fatty liver was common). 18989143
Chan-Tack KM, Struble KA, Birnkrant DB. Intracranial hemorrhage and liver-associated deaths associated with tipranavir/ritonavir: review of cases from the FDA's Adverse Event Reporting System. AIDS Patient Care STDS 2008; 22: 843-50. (Analysis of MedWatch reports on tipranavir with low dose ritonavir from 2005-2007 found 14 cases of intracerebral bleeding and 12 cases of liver related death [6 had HCV, 1 HBV coinfection]). 19025478
Burty C, Pavel S, Ghomari K, Vermersch A, Christian B, Pouaha J, Yazdanpanah Y, et al. Tolerability of fosamprenavir/ritonavir associated with zidovudine-lamivudine used as postexposure prophylaxis for HIV infection. J Acquir Immune Defic Syndr. 2008; 49: 334-6. (54 patients enrolled in a study of 4 weeks of zidovudine, lamivudine and fosamprenavir with low dose ritonavir for postexposure prophylaxis against acute HIV exposure; side effects were frequent, including nausea [73%], diarrhea [58%], fatigue [62%], rash [11%], but no "clinical or biological grade 3 or 4 event"; see Pavel, 2007). 18978479
Boffito M, Miralles D, Hill A. Pharmacokinetics, efficacy, and safety of darunavir/ritonavir 800/100 mg once-daily in treatment-naïve and -experienced patients. HIV Clin Trials 2008; 9: 418-27. (Review and comparison of efficacy and safety of once- vs twice-daily regimens of darunavir/ritonavir). 19203907
DeJesus E, Gottlieb MS, Gathe JC Jr, Greenberg ML, Guittari CJ, Zolopa AR. Safety and efficacy of enfuvirtide in combination with darunavir-ritonavir and an optimized background regimen in treatment-experienced human immunodeficiency virus-infected patients: the below the level of quantification study. Antimicrob Agents Chemother 2008; 52: 4315-9. (Among 137 patients with HIV receiving enfuvirtide with darunavir/ritonavir for 24 weeks there were 4 discontinuations and 18 serious adverse events, none were liver related and no mention of ALT elevations). 18809940
Vispo E. Warning on hepatotoxicity of darunavir. AIDS Rev 2008; 10: 63. (FDA released warning about clinical hepatotoxicity of darunavir boosted with low dose ritonavir in March 2008; during clinical development, hepatitis reported in 0.5% of recipients; several postmarketing reports of decompensation in patients with preexisting liver disease calls for careful monitoring). 18432296
Panther E, Thimme R, Blum HE. [Jaundice in an HIV-positive pregnant woman] Dtsch Med Wochenschr 2008; 133: 1560-2. German. (32 year old Nigerian woman with HIV infection on nelfinavir, zidovudine and lamivudine in last trimester of pregnancy developed jaundice [bilirubin 2.5 mg/dL, ALT 3126 U/L, Alk P 180 U/L]; further testing demonstrated anti-HEV positivity; antiretrovirals were restarted with resolution of the hepatitis; HEV tends to be severe in pregnant women). 18642217
Pineda JA, Pérez-Elí MJ, Peña JM, Luque I, Rodríguez-Alcantara F; Fosamprenavir Expanded Access Program Group. Low rate of adverse hepatic events associated with fosamprenavir/ritonavir-based antiretroviral regimens. HIV Clin Trials 2008; 9: 309-13. (Among 635 patients given fosamprenavir/ritonavir in an open access program, 3 developed ALT levels above 5 times ULN for a rate of 1% at 24 weeks; 2 with HCV and 1 with HBV; 4 patients with chronic hepatitis C had clinical decompensation and 1 died). 18977719
Soriano V, Puoti M, Garcia-Gascó P, Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN or ALT at lower levels if newly marketed agent; important to rule out other causes: problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Kumarasamy N, Venkatesh KK, Cecelia AJ, Devaleenal B, Lai AR, Saghayam S, Balakrishnan P, et al. Spectrum of adverse events after generic HAART in southern Indian HIV-infected patients. AIDS Patient Care STDS 2008; 22: 337-44. (Among 3154 patients with HIV infection treated with antiretroviral agents over a 4 year period at a single center in Southern India, hepatitis occurred in 3.5%, usually within the first 3 months; lactic acidosis was more common in women and was associated with stavudine use). 18422462
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirez and 4 miscellaneous combinations). 18955056
Molina JM, Andrade-Villanueva J, Echevarria J, Chetchotisakd P, Corral J, David N, Moyle G, et al.; CASTLE Study Team. Once-daily atazanavir/ritonavir versus twice-daily lopinavir/ritonavir, each in combination with tenofovir and emtricitabine, for management of antiretroviral-naive HIV-1-infected patients: 48 week efficacy and safety results of the CASTLE study. Lancet 2008; 372 (9639): 646-55. (Among 883 patients with HIV infection treated with atazanavir or lopinavir with ritonavir boost combined with tenofovir/emtricitabine, ALT elevations above 5 times ULN occurred in 1.8% vs 1.4% and bilirubin above 2.5 mg/dL in 34% vs 0.3%). 18722869
Macías J, Orihuela F, Rivero A, Viciana P, Márquez M, Portilla J, Ríos MJ, et al.; Hepatip Study Group. Hepatic safety of tipranavir plus ritonavir (TPV/r)-based antiretroviral combinations: effect of hepatitis virus co-infection and pre-existing fibrosis. J Antimicrob Chemother 2009; 63: 178-83. (Among 150 patients with HIV infection starting antiretroviral regimens including tipranavir/ritonavir, 12 [8%] developed ALT elevations above 5 times ULN: 7.5 per 100 patient-years). 18952618
Torti C, Lapadula G, Antinori A, Quirino T, Maserati R, Castelnuovo F, Maggiolo F, et al. Hyperbilirubinemia during atazanavir treatment in 2,404 patients in the Italian atazanavir expanded access program and MASTER cohorts. Infection 2009; 37: 244-9. (Among 2404 patients started on atazanavir [75% with low dose ritonavir boost], 45% developed bilirubin above 2.5 times ULN and 7.2% above 5 times ULN; risk factors being baseline bilirubin and ritonavir boost; bilirubin elevations were not associated with ALT elevations). 19471856
Jamois C, Riek M, Schmitt C. Potential hepatotoxicity of efavirenz and saquinavir/ritonavir coadministration in healthy volunteers. Arch Drug Inf 2009; 2: 1-7. (In a pharmacokinetic study done in healthy volunteers, one subject given saquinavir/ritonavir for 14 days developed abdominal pain and vomiting within 24 hours of adding efavirenz, with ALT rising to 145 U/L and then falling to normal 10 days after stopping medications; the study was terminated early). 19381337
Ingiliz P, Benhamou Y. Elevated liver enzymes in HIV monoinfected patients on HIV therapy: what are the implications? J HIV Ther 2009; 14: 3-7. (Review of the causes of serum enzyme elevations during antiretroviral therapy; nonnucleoside reverse transcriptase inhibitors are capable of causing a hypersensitivity reaction with liver injury arising during the first 6 weeks of therapy, as well as an immunologically mediated injury that arises 6-12 months after starting treatment; all protease inhibitors are metabolized in the liver by CYP 3A and have the potential to cause liver injury, this being most common with tipranavir). 19731558
Schmitt C, Riek M, Winters K, Schutz M, Grange S. Unexpected hepatotoxicity of rifampin and saquinavir/ritonavir in healthy male volunteers. Arch Drug Inf 2009; 2: 8-16. (In a phase I study of the combination of rifampin with saquinavir and ritonavir, 11 of 17 patients developed ALT elevations and gastrointestinal symptoms within 1-5 days of starting medication, with peak ALT levels of 400-5000 U/L, all resolving within 2 weeks of stopping). 19381336
Hughes CA, Robinson L, Tseng A, MacArthur RD. New antiretroviral drugs: a review of the efficacy, safety, pharmacokinetics, and resistance profile of tipranavir, darunavir, etravirine, rilpivirine, maraviroc, and raltegravir. Expert Opin Pharmacother 2009; 10: 2445-66. (Review of tipranavir, darunavir, etravirine, rilpivirine, maraviroc and raltegravir; regimens including tipranavir/ritonavir are associated with higher rates of significant ALT elevations [above 5 times ULN] than comparators; darunavir, the newest approved protease inhibitor, is an inhibitor of CYP 3A4, but pooled safety analyses showed no increased risk for adverse events vs comparator arms). 19678794
Bentué-Ferrer D, Arvieux C, Tribut O, Ruffault A, Bellissant E. Clinical pharmacology, efficacy and safety of atazanavir: a review. Expert Opin Drug Metab Toxicol 2009; 5: 1455-68. (Review of the chemistry, pharmacology, efficacy and safety of atazanavir; the most common "grade 2-4" side effect is dose dependent, reversible increase in indirect bilirubin, occurring in 20-60% of patients and more frequently with ritonavir boost; hyperbilirubinemia can be a reason for drug discontinuation, but largely for cosmetic reasons). 19863454
Haas DW, Koletar SL, Laughlin L, Kendall MA, Suckow C, Gerber JG, Zolopa AR, et al; A5213 StudyTeam. Hepatotoxicity and gastrointestinal intolerance when healthy volunteers taking rifampin add twice-daily atazanavir and ritonavir. J Acquir Immune Defic Syndr 2009; 50: 290-3. (In a small open label study assessing interactions of rifampin and atazanavir/ritonavir, the first 3 subjects who added protease inhibitors to rifampin developed nausea and ALT elevations within 24 hours [Peak ALT 792, 173 and 154 U/L] and study was stopped, values returning to normal within 1-2 weeks). 19194314
Ortu F, Weimer LE, Floridia M, Manconi PE. Raltegravir, tenofovir, and emtricitabine in an HIV-infected patient with HCV chronic hepatitis, NNRTI intolerance and protease inhibitors-induced severe liver toxicity. Eur J Med Res 2010; 15 (2): 81-3. (43 year old woman with HIV/HCV coinfection who developed symptomatic elevations of serum enzymes on saquinavir, fosamprenavir and again on darunavir, was adequately maintained on tenofovir/emtricitabine and raltegravir). 20452889
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (World wide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 cases, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen between 1997 and 2008 at a large hospital in Bangalore, India; none were attributed to antiretroviral agents). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir). 20949552
Heil EL, Townsend ML, Shipp K, Clarke A, Johnson MD. Incidence of severe hepatotoxicity related to antiretroviral therapy in HIV/HCV coinfected patients. AIDS Res Treat. 2010; 2010: 856542. (Among 56 patients with HIV-HCV coinfection who were started on antiretroviral therapy and followed at 2 infectious disesae clinics for an average of 3 years, 6 [11%] developed ALT or AST elevations above 5 times ULN, including 1 on indinavir, 1 saquinavir, 1 nelfinavir, but none on atazanavir or lopinavir). 21490905
Balayssac E, Autret-Leca E, Jonville-Béra AP, Diè-Kacou H, Beau-Salinas F. [Adverse reactions of atazanavir, fosamprenavir and tipranavir in "real life"]. Therapie 2010; 65: 121-8. (Summary of spontaneous reports of adverse side effects of HIV protease inhibitors to a French Pharmacovigilance Registry between 2004 and 2007, mentions hepatic adverse events from atazanavir [29 cases], fosamprenavir [5 cases] and tipranavir [5 cases], but most were hyperbilirubinemia alone [atazanavir] or serum enzyme elevations, often in patients with HIV-HCV coinfection). 20478244
Morsica G, Bianchi G, Bagaglio S, Conte C, Salpietro S, Porrino L, Uberti-Foppa C. Hepatic safety profile of darunavir with low-dose ritonavir (DRV/r) in HIV/HCV coinfected and HIV monoinfected patients. New Microbiol 2011; 34: 317-21. (Among 47 patients with HIV infection [18 coinfected with HCV] treated with darunavir/r for 72 weeks, median ALT and AST levels did not increase significantly and were never more than 1.6 times ULN). 21811753
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N: Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, none were attributed to an antiretroviral agent). 21788760
Kalyesubula R, Kagimu M, Opio KC, Kiguba R, Semitala CF, Schlech WF, Katabira ET. Hepatotoxicity from first line antiretroviral therapy: an experience from a resource limited setting. Afr Health Sci 2011; 11: 16-23. (Among 240 patients with HIV treated at a single center in Uganda, ALT elevations occurred in 4.2% by 14 weeks; few predictive features present except for antituberculosus therapy). 21572852
Merchante N, López-Cortés LF, Delgado-Fernández M, Ríos-Villegas MJ, Márquez-Solero M, Merino D, Pasquau J, et al; Grupo Andaluz para el Estudio de las Hepatitis Viricas (HEPAVIR) de la Sociedad Andaluza de Enfermedades Infecciosas (SAEI). Liver toxicity of antiretroviral combinations including fosamprenavir plus ritonavir 1400/100mg once daily in HIV/hepatitis C virus-coinfected patients. AIDS Patient Care STDS 2011; 25: 395-402. (Among 65 patients with HIV-HCV coinfection treated with an antiretroviral regimen including fosamprenavir/ritonavir for 48 weeks, 9 [14%] developed ALT elevations of above 5 times ULN, but none stopped therapy for this reason; neither cirrhosis nor fibrosis were associated with a higher likelihood of ALT elevations during therapy). 21688986
Dejesus E, Mills A, Bhatti L, Conner C, Storfer S. A randomised comparison of safety and efficacy of nevirapine vs. atazanavir/ritonavir combined with tenofovir/ emtricitabine in treatment-naïve patients. Int J Clin Pract 2011; 65: 1240-9. (Among 152 patients with HIV infection who were treated with nevirapine vs atazanavir/ritonavir, 1 patient in each group discontinued therapy for liver injury [enzyme elevations and jaundice]). 21999631
Daar ES, Tierney C, Fischl MA, Sax PE, Mollan K, Budhathoki C, Godfrey C, et al.; AIDS Clinical Trials Group Study A5202 Team. Atazanavir plus ritonavir or efavirenz as part of a 3-drug regimen for initial treatment of HIV-1. Ann Intern Med 2011; 154: 445-56. (Among 1848 patients with HIV infection treated with efavirenz or atazanavir/ritonavir in combination with nucleoside analogues, ALT elevations occurred in 2% and at a similar rate in both groups). 21320923
Minniear TD, Zeh C, Polle N, Masaba R, Peters PJ, Oyaro B, Akoth B, et al. Rash, hepatotoxicity and hyperbilirubinemia among Kenyan infants born to HIV-infected women receiving triple-antiretroviral drugs for the prevention of mother-to-child HIV transmission. Pediatr Infect Dis J 2012; 31: 1155-7. (Among 464 full term infants born to Kenyan mothers exposed to nevirapine or nelfinavir, there were no significant differences in rates of liver injury [0% vs 1.9%] or hyperbilirubinemia [3.9% vs 5.3%]). 22772167
Macías J, Neukam K, Mallolas J, López-Cortés LF, Cartón JA, Domingo P, Moreno S, et al.; COINS Study Team. Liver toxicity of initial antiretroviral drug regimens including two nucleoside analogs plus one non-nucleoside analog or one ritonavir-boosted protease inhibitor in HIV/HCV-coinfected patients. HIV Clin Trials 2012; 13: 61-9. (Retrospective analysis of 745 HIV infected patients started on antiviral regimens found ALT elevations above 5 times ULN in 11% starting nevirapine, 6% efavirenz, 10.5% protease inhibitor [PI]-based regimens, while discontinuations for enzyme elevations occurred in 13% on nevirapine, 4% efavirenz and 6% PI based regimens). 22510353
DeJesus E, Rockstroh JK, Henry K, Molina JM, Gathe J, Ramanathan S, Wei X, et al; GS-236-0103 Study Team. Co-formulated elvitegravir, cobicistat, emtricitabine, and tenofovir disoproxil fumarate versus ritonavir-boosted atazanavir plus co-formulated emtricitabine and tenofovir disoproxil fumarate for initial treatment of HIV-1 infection: a randomised, double-blind, phase 3, non-inferiority trial. Lancet 2012; 379 (9835): 2429-38. (Among 708 ppatients with HIV infection treated with boosted elvitegravir vs atazanavir based regimens for 48 weeks, HIV RNA response were similar and both regimens were "well tolerated", elevations in ALT occurring in 15% vs 22%, bilirubin 3% vs 96% which were severe in 0.5% vs 58%). 22748590
McDonald C, Uy J, Hu W, Wirtz V, Juethner S, Butcher D, McGrath D, et al. Clinical significance of hyperbilirubinemia among HIV-1-infected patients treated with atazanavir/ritonavir through 96 weeks in the CASTLE study. AIDS Patient Care STDS 2012; 26: 259-64. (Among 441 patients treated with atazanavir/r for 96 weeks in the CASTLE study [Molina 2008], 192 [44%] developed bilirubin elevations, among whom ALT elevations were no more frequent with in those without hyperbilirubinemia [4% vs 3%]; 3 patients discontinued therapy because of bilirubin elevations, but not because of concurrent ALT elevations). 22404426
Ha B, Wine B, Rodriguez-Alcantra F, Shaefer M. Hepatic safety profile of fosamprenavir-containing regimens in HIV-1-infected patients with or without hepatitis B or C coinfection. HIV Clin Trials 2012; 13: 171-7. (Among 1319 patients with HIV infection enrolled in clinical trials of fosamprenavir for at least 48 weeks, ALT elevations above 5 times ULN occurred in 14% of 205 patients with HBV or HCV coinfection, but only 1% of those with HIV monoinfection). 22592097
Surgers L, Lacombe K. Hepatoxicity of new antiretrovirals: a systematic review. Clin Res Hepatol Gastroenterol 2013; 37: 126-33. (Review of reports of heaptotoxicity of antiretroviral agents that had been recently approved including darunavir). 23522569
Wood R, Gathe JC, Givens N, Sedani S, Cheng K, Sievers J. Long-term safety study of fosamprenavir-containing regimens in HIV-1-infected patients. HIV Clin Trials 2013; 14:183-91. (Among 753 patients with HIV infection enrolled in long term extension studies of fosamprenavir containing regimens for up to 8 years, ALT elevations above 5 times ULN occurred in 8% overall, 3% of those with monoinfection and 13-35% of those with HBV or HCV coinfection; and among 5 deaths, none were due to liver disease). 24144895
Rockstroh JK, DeJesus E, Henry K, Molina JM, Gathe J, Ramanathan S, Wei X, et al; GS-236-0103 Study Team. A randomized, double-blind comparison of coformulated elvitegravir/cobicistat/emtricitabine/tenofovir DF vs ritonavir-boosted atazanavir plus coformulated emtricitabine and tenofovir DF for initial treatment of HIV-1 infection: analysis of week 96 results. J Acquir Immune Defic Syndr 2013; 62: 483-6. (Among 708 patients with HIV infection treated with evitegraveir/c vs atazanavir/r based regimens for up to 2 years, virologic response rates were similar while jaundice was reported in <1% vs 21% and led to discontinuation in 0% vs 0.6%; no mention of ALT elevations or clinically apparent liver injury). 23337366
Vispo E, Fernández-Montero JV, Labarga P, Barreiro P, Soriano V. Low risk of liver toxicity using the most recently approved antiretroviral agents but still increased in HIV-hepatitis C virus coinfected patients. AIDS 2013; 24; 27: 1187-8. (Among 1982 patients with HIV infection starting antiretroviral therapy, liver enzyme elevations occurred in 9% [17% with, 6% without HCV], but only 0.4% were greater than 5 times ULN [0.6% with and 0.2% without HCV]; rates were highest with darunavir and atazanavir and lowest with raltegravir and etravirine). 23739226
Samuel M, Bradshaw D, Perry M, Chan SY, Dhairyawan R, Byrne L, Smith K, et al. Antenatal atazanavir: a retrospective analysis of pregnancies exposed to atazanavir. Infect Dis Obstet Gynecol 2014; 2014: 961375. (Among 145 pregnancies in women with HIV infection treated with atazanavir, transient self-limited ALT or AST elevations occurred, but none required drug discontinuation, and there was no increase in frequency of neonatal hyperbilirubinemia over expected rates). 25328370
Floridia M, Ravizza M, Masuelli G, Giacomet V, Martinelli P, Degli Antoni A, Spinillo A, et al; Italian Group on Surveillance on Antiretroviral Treatment in Pregnancy. Atazanavir and lopinavir profile in pregnant women with HIV: tolerability, activity and pregnancy outcomes in an observational national study. J Antimicrob Chemother 2014; 69: 1377-84. (Among pregnancies in HIV positive women treated with lopinavir [n=322] or atazanavir [106] based regimens, there was no diferences in weight gain, glucose intolerance, but were higher median total cholesterol [239 vs 221 mg/dL] and triglycerides [226 vs 181 mg/dL] with lopinavir; no discontinuations for liver test abnormalities). 24370933
Di Biagio A, Nicolini LA, Lorenzini P, Puoti M, Antinori A, Cozzi-Lepri A, Gori A, et al, For The Icona Foundation Study Group. Liver enzyme elevation during darunavir-based antiretroviral treatment in HIV-1-infected patients with or without hepatitis C coinfection: data from the ICONA foundation cohort. HIV Clin Trials 2014; 15: 151-60. (Among 703 patients with HIV infection enrolled in an Italian multicenter registry who were treated with a darunavir/r based regimen, 101 [11 per 100 patient-years] developed liver test elevations, with a 3 fold higher risk among those with HCV coinfection). 25143024
Lapadula G, Costarelli S, Chatenoud L, Castelli F, Astuti N, Di Giambenedetto S, Quiros-Roldan E, et al; Italian MASTER Cohort. Risk of Liver Enzyme Elevation During Treatment With Ritonavir-Boosted Protease Inhibitors Among HIV-Monoinfected and HIV/HCV-Coinfected Patients. J Acquir Immune Defic Syndr 2015; 69: 312-8. (Among 6,193 patients with HIV infection who started antiretroviral therapy during follow up in a multicenter Italian registry, 761 [12%] had ALT or AST elevations above 5 times ULN, rates of elevations being higher among those with HIV-HCV coinfection than HIV infection alone [8 vs 1 per 100 patient-years]; multivariant analysis found no association of ALT elevations with specific protease inhibitor used). 25723139
Lê MP, Mandelbrot L, Descamps D, Soulié C, Ichou H, Bourgeois-Moine A, Damond F, et al. Pharmacokinetics, safety and efficacy of ritonavir-boosted atazanavir (300/100 mg once daily) in HIV-1-infected pregnant women. Antivir Ther 2015; 20: 507-13. (Among 103 women with HIV infection treated with atazanavir/r based regimens during pregnancy, there were no "clinical relevant" adverse events, only 1 woman with bilirubin above 2.5 mg/dL and 5 neonates with values above 5.8 mg/dL). 25599649
Rutstein RM, Samson P, Fenton T, Fletcher CV, Kiser JJ, Mofenson LM, Smith E, et al; PACTG 1020A Study Team. Long-term safety and efficacy of atazanavir-based therapy in HIV-infected infants, children and adolescents: the Pediatric AIDS Clinical Trials Group Protocol 1020A. Pediatr Infect Dis J 2015; 34: 162-7. (Among 195 children with HIV infection treated with atazanavir based regimens for 48 weeks, 9% developed bilirubin values above 5.1 mg/dL and 3% had ALT elevations above 2.5 times ULN). 25232777
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, 3 were attributed to antiretroviral agents [nevirapine, zidovudine and lamivudine], but none to HIV protease inhibitors). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 13 cases [1.5%] were attributed to antiretroviral therapy, including 3 to darunavir, 1 atazanavir and 1 nelfinavir). 25754159
Slama L, Landman R, Assoumou L, Benalycherif A, Samri A, Joly V, Pialoux G, et al; IMEA 040 DATA Study Group. Efficacy and safety of once-daily ritonavir-boosted atazanavir or darunavir in combination with a dual nucleos(t)ide analogue backbone in HIV-1-infected combined ART (cART)-naive patients with severe immunosuppression: a 48 week, non-comparative, randomized, multicentre trial (IMEA 040 DATA trial). J Antimicrob Chemother 2016; 71: 2252-61. (Among 120 patients with advanced AIDs treated with either atazanavir/r or darunavir/r based therapy for 48 weeks, 1 patient in both groups stopped therapy because of "hepatic cytolysis" and 1 on atazanavir for jaundice, but no details provided). 27068399
Cooper DA, Cordery DV, Zajdenverg R, Ruxrungtham K, Arastéh K, Bergmann F, Neto JL; study team. Tipranavir/Ritonavir (500/200 mg and 500/100 mg) was virologically non-iInferior to lopinavir/ritonavir (400/100 mg) at week 48 in trreatment-naïve HIV-1-infected patients: a randomized, multinational, multicenter trial. PLoS One 2016; 11: e0144917. (Among 558 treatment-naive patients with HIV infection treated with tipranavir/r [one of 2 dose of ritonavir] or lopinavir/r for 48 weeks, response rates were similar, but ALT elevations were more frequent with tipranavir [7%-22% vs 3.2%] which more frequently led to discontinuation [3%-7% vs 1%]). 26730818
Nasta P, Salmon D, d'Arminio Monforte A, Pimenta JM, Cerini C, Giralda M, Winnock M, et al. Fosamprenavir/ritonavir in patients with viral hepatitis coinfection: an observational multicohort study. HIV Clin Trials 2016; 17: 96-108. (Among 1096 patients with HIV infection treated with either fosamprenavir/r or lopinavir/r, ALT elevations above 200 U/L occurred in 5.6 per 100 person-years, and rates were similar for the two protease inhibitors). 27125364
Teófilo E, Rocha-Pereira N, Kuhlmann B, Antela A, Knechten H, Santos J, Jiménez-Expósito MJ; REMAIN study group. Long-term efficacy, tolerability, and renal safety of atazanavir/ritonavir-based antiretroviral therapy in a cohort of treatment-naïve patients with HIV-1 iInfection: the REMAIN Study. HIV Clin Trials 2016; 17: 17-28. (Among 517 patients with HIV infection treated with atazanavir/r based therapy and followed for 3 years, 16% discontinued therapy because of adverse events, 9% for hyperbilirubinemia). 26899539
Yunquera-Romero L, Asensi-Díez R, Del Rio-Valencia JC, Muñoz-Castillo I, Castaño-Carracedo MA. [Darunavir/cobicistat monotherapy. Experience in a tertiary hospital]. Rev Esp Quimioter 2016; 29: 308-317. (Among 78 patients with HIV infection who were switched from ritonavir to cobicistat to boost darunavir-based therapy, HCV RNA levels remained undetectable in 83% of patients and there were "no signficant differences" in serum ALT or AST levels with the change). 27888600
Antinori A, Meraviglia P, Monforte Ad, Castagna A, Mussini C, Bini T, Gianotti N, et al. Effectiveness, durability, and safety of darunavir/ritonavir in HIV-1-infected patients in routine clinical practice in Italy: a postauthorization noninterventional study. Drug Des Devel Ther 2016; 10: 1589-603. (Among 875 patients with HIV infection being treated with darunavir/r in an Italian clinical practice registry, darunavir was "effective and well tolerated", 2 patients discontinue therapy because of serum ALT elevations, but overall levels remained stable). 27226708
Pernas B, Grandal M, Tabernilla A, Cid P, Pértega S, Castro-Iglesias Á, Mena Á, et al. Long-term clinical experience with darunavir (2007-2015) in a large cohort of HIV-infected patients in Spain. J Med Virol 2016; 88: 2125-2131. (Among 173 patients with HIV infection who started antiretroviral therapy with darunavir between 2007 and 2015, 90% of patients had no "relevant" adverse events; no mention of ALT levels or liver related serious adverse events). 27218208
Kaspar MB, Sterling RK. Hyperbilirubinaemia in HIV-HCV co-infected patients on antiretroviral therapy: drug effect or liver disease severity? BMJ Open Gastroenterol 2016; 3: e000072. (Among 344 patients with HIV-HCV coinfection undergoing liver biopsy, 33% had hyperbilirubinemia; those attributable to indinavir [40%] or atazanavir [46%] did not correlate with hepatic fibrosis, whereas those elevations in patients on other antiretrovirals did correlate with biopsy fibrosis grade). 26966552
Fätkenheuer G, Jessen H, Stoehr A, Jung N, Jessen AB, Kümmerle T, Berger M, et al. PEPDar: A randomized prospective noninferiority study of ritonavir-boosted darunavir for HIV post-exposure prophylaxis. HIV Med 2016; 17: 453-9. (Among 305 patients with acute exposure to HIV who were treated with darunavir/r vs lopinavir/r based regimens for 28-30 days, none developed HIV infection and none suffered a serious adverse event; no mention of ALT elevations). 27166295
Masetti M, Magalotti D, Martino E, Andreone P, Scuteri A, Zoli M. A case of acute liver failure during ritonavir-boosted paritaprevir, ombitasvir and dasabuvir therapy in a patient with HCV genotype 1b cirrhosis. J Gastrointestin Liver Dis 2016; 25: 559-561. (84 year old man with HCV-related cirrhosis developed hepatic decompensation 13 days after starting Viekira Pak for HCV infection, with slow and incomplete recovery upon stopping). 27981315
Buzas C, Tantau M, Ciobanu L. Fatal acute liver failure during ritonavir-boosted paritaprevir, ombitasvir and dasabuvir plus ribavirin therapy. J Gastrointestin Liver Dis 2017; 26: 93-94. (65 year old woman with HCV related cirrhosis developed hepatic decompensation 3 days after starting Veikira Pak therapy for hepaittis C and died of hepatic failure 19 days later). 28338122
Fofiu C, Dobru D, Boeriu A. Potential pitfalls of Viekira Pak™ therapy in patients with HCV genotype 1b cirrhosis. J Gastrointestin Liver Dis 2017; 26: 94-95. (60 year old woman with HCV related cirrhosis developed decompensation 6 weeks after starting Viekira Pak for HCV infection [bilirubin rising from 2.1 to 6.8 mg/dL, INR 1.4 to 1.8], resolving slowly after discontinuation of the combination antiviral therapy; role of ritonavir unclear). 28338123
Menshawy A, Ismail A, Abushouk AI, Ahmed H, Menshawy E, Elmaraezy A, Gadelkarim M, et al. Efficacy and safety of atazanavir/ritonavir-based antiretroviral therapy for HIV-1 infected subjects: a systematic review and meta-analysis. Arch Virol 2017; 162: 2181-2190. (Systematic review of literature comparing atazanavir/r based regimens to darunavir/r or lopinavir/r, found rates of bilirubin elevations were markedly higher with atazanavir/r, but rates of ALT and AST elevations were similar). 28361290
Gallant JE, Koenig E, Andrade-Villanueva J, Chetchotisakd P, DeJesus E, Antunes F, Arastéh K, et al. Cobicistat versus ritonavir as a pharmacoenhancer of atazanavir plus emtricitabine/tenofovir disoproxil fumarate in treatment-naive HIV type 1-infected patients: week 48 results. J Infect Dis 2013; 208: 32-9. (Among 692 patients with HIV infection treated with atazanavir boosted with either ritonavir or cobicistat for 48 weeks, virologic response and adverse events rates were similar, but hyperbilirubinemia was more frequent with cobicistat [65% vs 57%] as were ALT elevations above 5 times ULN [3.2% vs 2.0%], but there were no drug related serious hepatic adverse events). 23532097